# Infliximab

## OVERVIEW

### Introduction

Infliximab is a monoclonal antibody to human tumor necrosis factor alpha (TNFα) which has potent antiinflammatory activity and is used in the therapy of severe inflammatory bowel disease and rheumatoid arthritis. Infliximab has been linked to many instances of idiosyncratic acute liver injury and is a well known cause of reactivation of hepatitis B.

### Background

Infliximab (in flix' i mab) is a mouse-human chimeric monoclonal antibody to TNFα which binds avidly to serum and tissue bound TNFα, causing its inactivation and degradation. Inhibition of TNFα activity leads to modulation of the inflammatory and pain pathways activated by this cytokine. Infliximab was approved for use in the United States in 1998 and current indications include rheumatoid arthritis, ankylosing spondylitis, psoriatic arthritis and severe psoriasis, Crohn disease (adult and pediatric) and ulcerative colitis (adult and pediatric). Infliximab is considered a disease modifying antirheumatic drug (DMARD) and has been shown to improve symptoms as well as joint and cartilage damage in the inflammatory arthritidies. Infliximab is available in vials containing 100 mg under the brand name of Remicade. The dose of infliximab varies by indication (3 to 10 mg/kg per intravenous infusion), and it is generally given at 0, 2 and 6 weeks, and then in a maintenance dose at 8 week intervals. Common side effects include infusion reactions, upper respiratory infections, headache, abdominal pain, rash and fever. Rare but potentially severe side effects include severe infections, fungal infections, seizures, heart failure, renal failure, bone marrow suppression, demyelinating diseases, lupus-like syndrome, hepatic injury, increased risk of lymphoma and other malignancies, hypersensitivity reactions, and Stevens Johnson syndrome. TNFα antagonists are also capable of causing immune suppression, resulting in reactivation of tuberculosis and hepatitis B.

### Hepatotoxicity

Infliximab has been associated with at least four forms of hepatic injury which have quite separate causes and different clinical outcomes. First, infliximab can cause serum aminotransferase elevations, which generally arise after 2 to 5 infusions. These elevations can be transient and are usually asymptomatic, but in some instances they become progressively higher with each infusion necessitating discontinuation (Case 2). Serum alkaline phosphatase levels may also rise, but generally to a lesser degree. Progression to symptomatic hepatitis with jaundice can also occur, but the liver test abnormalities usually resolve within 4 to 12 weeks of stopping treatment. Patients with this form of infliximab hepatotoxicity usually tolerate etanercept without similar problems.

A second type of liver injury associated with infliximab use is a hepatocellular injury typically associated with autoimmune markers. Infliximab induces autoantibodies including antinuclear (ANA), smooth muscle (SMA) and double-stranded DNA autoantibodies (anti-dsDNA), in a high proportion of patients. These autoantibodies are usually not accompanied by clinically apparent autoimmune conditions. In rare instances, however, a lupus-like syndrome or frank autoimmune hepatitis accompanies these autoantibodies. These complications generally arise after 6 or more months of therapy and are usually symptomatic, although the course is often anicteric and mild. The autoimmune hepatitis is marked by a hepatocellular pattern of serum enzyme elevations and frequently the presence of ANA or other autoantibodies. Liver biopsy usually shows changes typical of autoimmune hepatitis, such as interface hepatitis, focal liver cell necrosis and intense mononuclear cell infiltrates that may include plasma cells. The liver injury usually improves upon stopping infliximab and starting corticosteroids, but can be severe and lead to death or need for emergency liver transplant.

A third form of Infliximab induced liver injury is a cholestatic form of liver injury that can arise as early as a few days to up to 24 weeks after starting therapy. Symptoms include jaundice and pruritus, and liver biopsy shows cholestasis with mild inflammation. The course can be prolonged, but is usually self-limiting (Case 1). Autoantibodies and immunoallergic features are typically not present.

A fourth type of hepatic injury caused by infliximab is reactivation of chronic hepatitis B (Case 3). Patients receiving infliximab for an autoimmune condition who are also HBsAg carriers can have a reactivation of hepatitis B virus (HBV) activity with rise in serum HBV DNA concentrations, followed by abnormal ALT levels and clinically apparent hepatitis with jaundice. Reactivation of hepatitis B can be severe and the mortality rate among jaundiced cases is at least 10%. The rise in HBV DNA levels usually occurs within the first few months of infliximab therapy, but is clinically silent until after ALT levels rise 2 to 6 months later. Antiviral agents with potent activity against HBV such as entecavir or tenofovir appears to prevent reactivation of hepatitis B, and early intervention (before onset of symptoms) with antivirals may ameliorate the course of illness. Much more rarely, reactivation occurs in patients with anti-HBc without HBsAg (serologic pattern of previous HBV infection). In such patients, careful monitoring with testing for HBV DNA at regular intervals may be used instead of prophylaxis. Appearance of HBV DNA in serum during therapy should lead to prompt initiation of antiviral therapy. The anti-TNF inhibitors have little or no effects on hepatitis C virus levels and have been safely used in patients with chronic hepatitis C as well as with other serious chronic liver diseases such as alcoholic liver disease, nonalcoholic fatty liver disease and primary biliary cirrhosis.

Likelihood score: A (well established cause of clinically apparent liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury caused by infliximab is probably due to autoimmunity caused by the immunomodulatory therapy. While a high proportion of patients develop autoantibodies either de novo or in rising titer, only rare persons develop clinically apparent autoimmune conditions, such as lupus-like syndrome or autoimmune hepatitis. The cholestatic forms of injury may have a different pathogenesis. Because infliximab is a monoclonal antibody, it is not metabolized by the liver except as is typical for most proteins.

### Outcome and Management

The liver injury caused by infliximab is usually mild and rapidly reversed once therapy is stopped. However, fatal instances of HBV reactivation and induction of autoimmune hepatitis due to infliximab have been reported, and regular monitoring of patients early during the course of infliximab is recommended. Patients who are to start infliximab therapy should be screened for evidence of hepatitis B, and those with preexisting HBsAg should be offered prophylaxis with an oral antiviral agent such as tenofovir or entecavir. Patients who develop an autoimmune hepatitis-like syndrome during infliximab therapy may not recover promptly with stopping the TNFα antagonist and may require corticosteroid therapy. In this event, the dose of the corticosteroid should be kept to a minimum to control the disease and, ultimately, attempts should be made to withdraw immune suppression (or decrease to levels used before administration of infliximab). Rechallenge with infliximab is not recommended after liver injury with symptoms or jaundice, but there does not appear to be cross reactivity in hepatic injury between infliximab and other TNFα antagonists especially etanercept, which is not a monoclonal antibody but rather a modified form of the TNFα receptor.

Drug Class: Antirheumatic Agents; Dermatologic Agents; Gastrointestinal Agents, Inflammatory Bowel Disease Agents

Other Drugs in the Subclass, Tumor Necrosis Factor Antagonists: Adalimumab, Certolizumab [underlined: Pegol], Etanercept, Golimumab

## CASE REPORTS

### Case 1. Cholestatic hepatitis associated with infliximab therapy.(1)

A 44 year old woman with long standing Crohn disease on a regimen of mesalamine, mercaptopurine (150 mg/day) and prednisone (10 mg/day) was started on infliximab (5 mg/kg infusions). 19 days after the initial infusion she developed fatigue, anorexia and nausea, followed a few days later by dark urine, jaundice and pruritus. Evaluation demonstrated jaundice without fever, rash or signs of chronic liver disease. She denied risk factors for viral hepatitis and excessive alcohol use. She was taking no over-the-counter or herbal medications. She had modest elevations in serum aminotransferase levels (ALT 149 U/L, AST 119 U/L), no elevation in alkaline phosphatase (55 U/L), but marked elevation in gamma glutamyl transpeptidase (GGT) with an initial bilirubin was 7.4 mg/dL (Table). She had no eosinophilia. Tests for hepatitis A, B and C were negative and autoantibodies were negative except for a weakly positive antinuclear antibody. She continued to worsen over the ensuing week. Ultrasound of the abdomen was unrevealing, and retrograde cholangiopancreatography was normal. A liver biopsy showed bland cholestasis with minimal inflammation and no fibrosis. With conservative management, she improved and two months after initial presentation her liver tests had returned to normal. She continued her chronic regimen of mercaptopurine and prednisone.

#### Key Points

Medication: | Infliximab (single infusion of 5 mg/kg)
Pattern: | Mixed (R=3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 19 days
Recovery: | 2 months
Other medications: | Chronically, mercaptopurine, prednisone, mesalamine, folic acid and oral contraceptives (for many years)

#### Laboratory Values

Time After Infusion | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 38 | 57 | 1.0 | Before infusion
21 days | 119 | 55 | 7.4
23 days | 163 | 65 | 12.3 | GGT 581 U/L
26 days | 223 | 301 | 19.2 | ERCP normal
28 days | 153 | 261 | 16.8 | Liver biopsy
32 days | 104 | 282 | 13.8
12 weeks | 13 | 56 | 1.1
Normal | <40 | <213 | <1.2

#### Comment

An early report documenting a cholestatic hepatitis arising 19 days after an initial infusion of infliximab. The hepatitis was not accompanied by appearance of autoantibodies and there was no evidence for reactivation of an underlying hepatitis. The liver biopsy was characterized by a bland cholestasis. In the absence of exposures to other potential causes of drug induced liver injury, it is difficult to ascribe this episode to anything except infliximab. Nevertheless, the time to onset, pattern of presentation and course, while being typical of drug induced liver injury, are atypical of the hepatotoxicity of infliximab and more typical of mercaptopurine. The concurrent use of prednisone and mercaptopurine may have altered the clinical course; both agents were continued.

### Case 2. Serum aminotransferase elevations following infliximab therapy.(2)

A 48 year old man with long standing, symptomatic ankylosing spondylitis was started on infliximab (5 mg/kg) infusions which were planned to be given at 0, 2 and 6 weeks, followed by every 8 weeks thereafter. The infusions were followed by marked improvement in his clinical symptoms and inflammatory markers. Serum aminotransferase levels, which had been normal before therapy, were slightly elevated after the second infusion and rose even higher after the third and fourth (Table). He remained asymptomatic and anicteric without rash, fever or signs of hepatic disease. Tests for hepatitis A, B and C were negative as were serum autoantibodies. An abdominal ultrasound showed no abnormalities. He denied significant alcohol intake. Other medications included nonsteroidal antiinflammatory agents only, which had been discontinued early. Once his serum aminotransferase levels rose above 10 times the upper limit of normal (week 22), the infliximab infusions were stopped, and he was monitored on no therapy. ALT levels fell to normal within 10 weeks, and he was started on etanercept infusions (25 mg twice weekly), which led to a prompt clinical response and serum enzymes remained normal during the subsequent 20 weeks of treatment.

#### Key Points

Medication: | Infliximab (4 infusions of 5 mg/kg)
Pattern: | Hepatocellular (R=8.2)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 6 weeks
Recovery: | 10 weeks after stopping
Other medications: | Flogoprofen (NSAID)

#### Laboratory Values

Time after first infusion | Time after stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | | 35
0 | | 32 | 32 | Normal | First infusion
2 weeks | | 35 | | | Second infusion
6 weeks | | 60 | | | Third infusion
14 weeks | | 382 | 88 | 0.6 | Fourth infusion
22 weeks | 0 | 656 | 140 | | Infliximab stopped
26 weeks | 4 weeks | 370
32 weeks | 10 weeks | | 45 | Normal | Etanercept started
38 weeks | 4 months | 35 | Normal
44 weeks | 5 months | | 30 | Normal
1 year | 6 months | 25 | Normal
Normal | | <45 | <50 | <1.2

* Some values are estimated from Figure 1.

#### Comment

This patient developed serum aminotransferase elevations without jaundice or symptoms starting after 2 infusions of infliximab, leading to its discontinuation after 4 infusions when ALT levels were greater than 10-fold elevated. The patient had had an excellent clinical response to infliximab and was switched to etanercept, a non-monoclonal antibody based TNFa blocker, which yielded a similar clinical response without ALT elevations. The cause of the ALT elevations during infliximab therapy is not known, but in this situation it did not appear to be immunologically mediated.

### Case 3. Reactivation of hepatitis B during infliximab therapy.(3)

A 43 year old woman with Crohn disease and the HBsAg carrier state who had been treated unsuccessfully with corticosteroids and sulfasalazine was started on intravenous infliximab in a regimen of 5 mg/kg at 0, 2 and 6 weeks, followed by repeat infusions every 8 weeks. After the third infusion, mercaptopurine was added. She was known to be HBsAg-positive for several years, but was asymptomatic of liver disease and had always had normal serum aminotransferase levels as well as absence of HBeAg, and no or only low levels of HBV DNA in serum. After the fourth infusion of infliximab, however, her HBV DNA and ALT levels began to rise and lamivudine (100 mg daily) was started (Table). After the sixth infusion when HBV ALT levels reached 5 times the upper limit of normal, infliximab, sulfasalazine and mercaptopurine were stopped. Despite lamivudine therapy, HBV DNA levels subsequently rose to >10 million copies/mL and ALT peaked at 350 U/L. A liver biopsy showed moderate chronic hepatitis and mild fibrosis. She began to improve thereafter and lamivudine was continued. Three months later, serum aminotransferase levels were again normal and HBV DNA was undetectable, but her Crohn disease was again active. Infliximab was restarted, but she had no further evidence of reactivation of hepatitis B.

#### Key Points

Medication: | Infliximab (6 infusions of 5 mg/kg)
Pattern: | Probably hepatocellular (alkaline phosphatase levels not provided)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 4-5 months
Recovery: | 3-4 months after stopping
Other medications: | Mercaptopurine, sulfasalazine, lamivudine

#### Laboratory Values

Time after first infusion | Infliximab Infusions | ALT* (U/L) | HBV DNA* (copies/mL) | Other
Pre | 0 | 15 | <2000
1 month | 2 | 25 | <2000
2 months | 3 | 40 | 300,000 | Lamivudine started
4 months | 4 | 38 | 200,000
6 months | 5 | 57 | 200,000
8 months | 6 | 60 | 1,200,000
8.5 months | | 145 | 20,000,000 | Infliximab held
9 months | | 239 | 300,000
9.5 months | | 320 | 10,000
9.7 months | | 245 | 4,000
10 months | 7 | 19 | <100 | Infliximab restarted
1 year | 8 | 15 | <100
1.3 years | 9 | 11 | <100
Normal | | <50 | None

* Some values are estimated from Figure 1.

#### Comment

This patient had a mild episode of reactivation of hepatitis B (without jaundice or hepatic decompensation) while being treated with infliximab for Crohn disease. The timing of onset of reactivation is typically after 1 to 4 months of treatment. Initially, HBV DNA levels rise and, 1 to 2 months later, ALT levels increase and symptoms and jaundice may arise. This patient’s relatively mild course may have been due to the fact that lamivudine was started promptly when HBV DNA levels rose. While lamivudine is a potent inhibitor of HBV replication, it generally requires 1 to 3 months of therapy before its full effects are present. Thus, starting lamivudine after reactivation has begun is often not successful. Most studies of immune suppression in HBsAg carriers have shown that prophylaxis is more effective than early intervention. Once lamivudine had been given for several months, the patient was able to tolerate infliximab without further evidence of reactivation. The lamivudine, however, should be continued.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Infliximab – Remicade®

DRUG CLASS

Antirheumatic Agents; Dermatologic Agents; Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=infliximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Infliximab | 170277-31-3 | Monoclonal antibody

## CITED REFERENCES

1 Menghini VV, Arora AS. Infliximab-associated reversible cholestatic liver disease. Mayo Clin Proc 2001; 76: 84-6. 11155419
2 García Aparicio AM, Rey JR, Sanz AH, Alvarez JS. Successful treatment with etanercept in a patient with hepatotoxicity closely related to infliximab. Clin Rheumatol 2007; 26: 811-3. 16550301
3 Ojiro K, Naganuma M, Ebinuma H, Kunimoto H, Tada S, Ogata H, Iwao Y, et al. Reactivation of hepatitis B in a patient with Crohn's disease treated using infliximab. J Gastroenterol 2008; 43: 397-401. 18592158

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2026

Abbreviations Used: TNF, tumor necrosis factor alpha; anti-TNF, antibody to TNF; ANA, anti-nuclear antigen; dsDNA, double stranded DNA; HBV, hepatitis B virus; HBsAg, hepatitis B surface antigen; anti-HBs, antibody to HBsAg; anti-HBc, antibody to hepatitis B core antigen; HBeAg, hepatitis B e antigen; anti-HBe, antibody to HBeAg; HCV, hepatitis C virus, anti-HCV, antibody to HCV.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; no mention of infliximab or other anti-tumor necrosis factor (anti-TNF) agents).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents published in 2013; all of the monoclonal anti-TNF agents have been linked to cases of hepatoxicity ranging in severity from asymptomatic aminotransferase elevations to acute liver failure).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Maini R, St Clair EW, Breedveld F, Furst D, Kalden J, Weisman M, Smolen J, et al. Infliximab (chimeric anti-tumour necrosis factor alpha monoclonal antibody) versus placebo in rheumatoid arthritis patients receiving concomitant methotrexate: a randomised phase III trial. ATTRACT Study Group. Lancet 1999; 354: 1932-9. (Controlled trial of infliximab vs placebo for 30 weeks in 428 patients with rheumatoid arthritis receiving methotrexate, found no difference in rates of ALT elevations between the two groups [37% vs 29%] and no cases of clinically apparent liver injury). 10622295
Menghini VV, Arora AS. Infliximab-associated reversible cholestatic liver disease. Mayo Clin Proc 2001; 76: 84-6. (44 year old woman with Crohn disease developed fatigue 19 days after single infusion of infliximab with subsequent jaundice [bilirubin 7.4 rising to 19.2 mg/dL, Alk P 55 U/L, ALT 149 U/L], liver biopsy showed bland cholestasis, ANA was weakly positive; abnormalities resolved in 2 months: Case 1). 11155419
Saleem G, Li SC, MacPherson BR, Cooper SM. Hepatitis with interface inflammation and IgG, IgM, and IgA anti-double-stranded DNA antibodies following infliximab therapy: comment on the article by Charles et al. Arthritis Rheum 2001; 44: 1966-8. (36 year old woman with rheumatoid arthritis developed symptoms shortly after third monthly infusion of infliximab with subsequent jaundice [bilirubin 16.6 mg/dL, ALT 448 U/L] and increase in ANA titer [1:160] with IgG antibodies to dsDNA, improving rapidly with prednisone therapy). 11508453
Biancone L, Pavia M, De Vecchio Blanco G, D'Inca R, Castiglione F, De Nigris F, Doldo P, et al. Hepatitis B and C virus infection in Crohn's disease. Inflamm Bowel Dis 2001; 7: 287-94. (Among 332 Italian patients with Crohn disease, 7.4% had anti-HCV and 2.1% HBsAg compared to 5.1% and 2.1% of Italian controls; no clear change in hepatitis with therapy of Crohn disease in small numbers of cases studied retrospectively). 11720317
Day R. Adverse reactions to TNF-alpha inhibitors in rheumatoid arthritis. Lancet 2002; 359: 540-1. (Editorial on the severe side effects of long term anti-TNF therapy in rheumatoid arthritis focusing upon reactivation of tuberculosis, induction of a lupus-like syndrome and rare instances of cancer; no mention of hepatotoxicity). 11867103
Hanauer SB, Feagan BG, Lichtenstein GR, Mayer LF, Schreiber S, Colombel JF, Rachmilewitz D, et al.; ACCENT I Study Group. Maintenance infliximab for Crohn's disease: the ACCENT I randomised trial. Lancet 2002; 359: 1541-9. (Randomized trial of infliximab vs placebo in 573 patients with Crohn disease; no mention of hepatotoxicity). 12047962
Biancone L, Del Vecchio Blanco G, Pallone F, Castiglione F, Bresci G,Sturniolo G; Italian Group for the Study of the Colon and Rectum. Immunomodulatory drugs in Crohn's disease patients with hepatitis B or C virus infection. Gastroenterology 2002; 122: 593-4. (Further analysis of 4 patients with Crohn disease and hepatitis B who received immunomodulatory medications; no instances of reactivation). 11845808
Michel M, Duvoux C, Hezode C, Cherqui D. Fulminant hepatitis after infliximab in a patient with hepatitis B virus treated for an adult onset Still's disease. J Rheumatol 2003; 30: 1624-5. (Patients with adult Still disease and HBsAg [without HBeAg or HBV DNA] developed fever, rash and severe hepatitis after a second infusion of infliximab [direct bilirubin 14.6 mg/dL, ALT 30 times ULN], progressing to acute liver failure and liver transplant but without detectable HBV DNA; no testing for delta hepatitis). 12858469
Ostuni P, Botsios C, Punzi L, Sfriso P, Todesco S. Hepatitis B reactivation in a chronic hepatitis B surface antigen carrier with rheumatoid arthritis treated with infliximab and low dose methotrexate. Ann Rheum Dis 2003; 62: 686-7. (59 year old man with rheumatoid arthritis and HBsAg in serum developed hepatitis 18 months after starting infliximab [bilirubin 1.3 mg/dL, ALT 573 U/L] with presence of IgM anti-HBc and increase in serum HBV DNA polymerase activity; resolution in 2 months). 12810441
Peterson JR, Hsu FC, Simkin PA, Wener MH. Effect of tumour necrosis factor alpha antagonists on serum transaminases and viraemia in patients with rheumatoid arthritis and chronic hepatitis C infection. Ann Rheum Dis 2003; 62: 1078-82. (Monitoring of 24 patients with both rheumatoid arthritis and hepatitis C found no overall changes in ALT, AST, Alk P or HCV RNA levels during therapy with etanercept or infliximab over a period of 2-34 months). 14583571
Furst DE, Schiff MH, Fleischmann RM, Strand V, Birbara CA, Compagnone D, Fischkoff SA, et al. Adalimumab, a fully human anti tumor necrosis factor-alpha monoclonal antibody, and concomitant standard antirheumatic therapy for the treatment of rheumatoid arthritis: results of STAR (Safety Trial of Adalimumab in Rheumatoid Arthritis). J Rheumatol 2003; 30: 2563-71. (Controlled trial of 24 weeks of adalimumab vs placebo in 636 patients with rheumatoid arthritis; adverse events were similar between the two groups with no differences in mean ALT or AST levels; adalimumab group had higher rates of de novo autoantibody formation [ANA 27% vs 15%, anti-DNA 13% vs 1%]). 14719195
Weinblatt ME, Keystone EC, Furst DE, Moreland LW, Weisman MH, Birbara CA, Teoh LA, et al. Adalimumab, a fully human anti-tumor necrosis factor alpha monoclonal antibody, for the treatment of rheumatoid arthritis in patients taking concomitant methotrexate: the ARMADA trial. Arthritis Rheum 2003; 48: 35-45. (Controlled trial of 24 weeks of adalimumab vs placebo in 271 patients with rheumatoid arthritis found no significant changes in serum ALT levels and no instance of clinically apparent liver injury). 12528101
Khanna D, McMahon M, Furst DE. Safety of tumour necrosis factor-alpha antagonists. Drug Saf 2004; 27: 307-24. (Review of safety of anti-TNF agents based on literature and FDA reports found no evidence of worsening of hepatitis C during therapy, but there was a chance of reactivation of hepatitis B, at least by infliximab; no discussion of hepatotoxicity). 15061685
Oniankitan O, Cuvoux C, Challine D, Mallat A, Chevalier X, Pawlotsky J-M, Claudepierre P. Infliximab therapy for rheumatic diseases in patients with chronic hepatitis B or C. J Rheumatol 2004; 31: 107-9. (Two patients with rheumatoid arthritis treated for one year with infliximab had no worsening of liver disease; one with hepatitis B was on lamivudine, one with hepatitis C had no change in HCV RNA levels). 14705228
Esteve M, Saro C, Gonzalez-Huix F, Suarez F, Fone M, Viver JM. Chronic hepatitis B reactivation following infliximab therapy in Crohn's disease patients: need for primary prophylaxis. Gut 2004; 53: 1363-5. (Among 3 patients with hepatitis B and Crohn disease, 2 developed a severe flare of hepatitis B after 2-3 months of infliximab therapy; the patient who did not suffer reactivation was being treated with lamivudine). 15306601
Parke FA, Reveille JD. Anti-tumor necrosis factor agents for rheumatoid arthritis in the setting of chronic hepatitis C infection. Arthritis Rheum 2004; 51: 800-4. (Among 5 patients with rheumatoid arthritis and HCV infection who were treated with etanercept or infliximab for 8-49 months, none had worsening of serum ALT levels and HCV RNA levels were stable or decreased). 15478165
Feletar M, Brockbank JE, Schentag CT, Lapp V, Gladman DD. Treatment of refractory psoriatic arthritis with infliximab: a 12 month observational study of 16 patients. Ann Rheum Dis 2004; 63: 156-61. (Among 16 patients with psoriasis treated with infliximab, 3 developed asymptomatic ALT elevations [141, 434 and 150 U/L], leading to early discontinuation; all resolved rapidly, 2 were on methotrexate). 14722204
Magliocco MA, Gottlieb AB. Etanercept therapy for patients with psoriatic arthritis and concurrent hepatitis C virus infection: report of 3 cases. J Am Acad Dermatol 2004; 51: 580-4. (Three men, ages 51-54 years, with psoriasis and chronic hepatitis C received etanercept for 3-7 months with no change in serum ALT or AST levels and slight decrease in HCV RNA levels in two). 15389194
Calabrese LH, Zein N, Vassilopoulos D. Safety of antitumour necrosis factor(anti-TNF) therapy in patients with chronic viral infections: hepatitis C, hepatitis B, and HIV infection. Ann Rheum Dis 2004; 63 Suppl 2: ii18-ii24. (Review of the safety and complications of anti-TNF therapy in patients with concurrent hepatitis B or C or HIV infection). 15479865
Eriksson C, Engstrand S, Sundqvist KG, Rantapää-Dahlqvist S. Autoantibody formation in patients with rheumatoid arthritis treated with anti-TNF alpha. Ann Rheum Dis 2005; 64: 403-7. (Among 53 patients with rheumatoid arthritis treated with infliximab, ANA titers frequently increased and a proportion of patients developed anti-dsDNA while symptoms improved and rheumatoid factor titers fell). 15297281
Anelli MG, Torres DD, Manno C, Scioscia C, Iannone F, Covelli M, Schena FP, et al. Improvement of renal function and disappearance of hepatitis B virus DNA in a patient with rheumatoid arthritis and renal amyloidosis following treatment with infliximab. Arthritis Rheum 2005; 52: 2519-20. (36 year old woman with rheumatoid arthritis, amyloidosis with presence of HBsAg and anti-HDV in serum was treated successfully with infliximab without reactivation, despite lack of antiviral prophylaxis; serum ALT levels, however rose perhaps due to worsening of delta hepatitis). 16052569
Germano V, Picchianti Diamanti A, Baccano G, Natale E, Onetti Muda A, Priori R, Valesini G. Autoimmune hepatitis associated with infliximab in a patient with psoriatic arthritis. Ann Rheum Dis 2005; 64: 1519-20. (53 year old woman with psoriasis developed persistent ALT elevations after 6 infusions of infliximab [ALT 234 U/L], with rise in antinuclear and anti-smooth muscle antibodies, liver biopsy showing chronic hepatitis and mild fibrosis, improving with stopping infliximab). 16162908
Infliximab: lymphomas and severe hepatitis. Prescrire Int 2005; 14: 179. (FDA reported 35 cases of severe liver damage due to infliximab including fatal cases of acute liver failure, autoimmune hepatitis and exacerbations of chronic hepatitis B). 16285074
Magro F, Pereira P, Carneiro F, Veloso FT. Reactive hepatitis in a patient with Crohn's disease successfully treated with infliximab: does tumor necrosis factor alpha play a role in reactive hepatitis? Inflamm Bowel Dis 2005; 11: 88-90. (21 year old woman with Crohn disease had elevations in ALT [198 U/L] and Alk P [440 U/L], which improved after infliximab therapy and correlated with disease activity). 15674127
Mizuta M, Schuster MG. Cytomegalovirus hepatitis associated with use of anti-tumor necrosis factor-alpha antibody. Clin Infect Dis 2005; 40: 1071-2. (45 year old woman with Crohn disease developed fever and abnormal liver tests [ALT 282 U/L, Alk P 845 U/L, bilirubin 1.1 mg/dL], and liver biopsy showing changes of cytomegalovirus hepatitis, resolving rapidly with ganciclovir therapy). 15825012
Wendling D, Auge B, Bettinger D, Lohse A, Le Huede G, Bresson-Hadni S, Toussirot E, et al. Reactivation of a latent precore mutant hepatitis B virus related chronic hepatitis during infliximab treatment for severe spondyloarthropathy. Ann Rheum Dis 2005; 64: 788-9. (35 year old woman with HBsAg [normal ALT levels and no HBeAg] and ankylosing spondylitis developed rising levels of HBV DNA followed by ALT elevations after starting infliximab therapy and improved on lamivudine therapy). 15834064
Zein NN; Etanercept Study Group. Etanercept as an adjuvant to interferon and ribavirin in treatment-naive patients with chronic hepatitis C virus infection: a phase 2 randomized, double-blind, placebo-controlled study. J Hepatol 2005; 42: 315-22. (Controlled trial of adding etanercept to interferon and ribavirin therapy of chronic hepatitis C found similar rates of sustained response [32% vs 42%] and no evidence of worsening of hepatitis during etanercept therapy). 15791697
Ueno Y, Tanaka S, Shimamoto M, Miyanaka Y, Hiyama T, Ito M, Kitadai Y, et al. Infliximab therapy for Crohn's disease in a patient with chronic hepatitis B. Dig Dis Sci 2005; 50: 163-6. (19 year old woman with Crohn disease and HBsAg, developed rise in HBV DNA levels followed by ALT increase after starting infliximab, resolving within 2 months of stopping, without antiviral therapy). 15712655
Scheinfeld N. Adalimumab: a review of side effects. Expert Opin Drug Saf 2005; 4: 637-41. (Review of side effects of adalimumab therapy mentions that it can induce a lupus-like syndrome [~0.1%] and minor ALT elevations). 16011443
Schreiber S, Rutgeerts P, Fedorak RN, Khaliq-Kareemi M, Kamm MA, Boivin M, Bernstein CN, et al.; CDP870 Crohn's Disease Study Group. A randomized, placebo-controlled trial of certolizumab pegol (CDP870) for treatment of Crohn's disease. Gastroenterology 2005; 129: 807-18. (Preliminary results of a controlled trial of certolizumab in 292 patients with Crohn disease; "Serial hematologic and biochemical measurements did not show the treatment to have any untoward events"). 16143120
Kaushik VV, Moots RJ. CDP-870 (certolizumab) in rheumatoid arthritis. Expert Opin Biol Ther 2005; 5: 601-6. (Review of safety and efficacy of certolizumab in rheumatoid arthritis; no serious side effects reported and no mention of hepatotoxicity). 15934837
Bratcher JM, Korelitz BI. Toxicity of infliximab in the course of treatment of Crohn's disease. Expert Opin Drug Saf 2006; 5: 9-16. (Review of safety of infliximab for Crohn disease; postmarketing reports of occasional cases of acute liver failure, jaundice, autoimmune hepatitis and cholestasis; single case report of cholestatic hepatitis). 16370952
Desai SB, Furst DE. Problems encountered during anti-tumour necrosis factor therapy. Best Pract Res Clin Rheumatol 2006; 20: 757-90. (Extensive review of side effects of use of anti-TNF blockers; in 7 reports on 29 patients with hepatitis C, no flares of disease occurred on infliximab or etanercept; 11 report cases of use in hepatitis B with at least 3 instances of reactivation, one fatal, largely with infliximab and methotrexate). 16979537
Ierardi E, Della Valle N, Nacchiero MC, De Francesco V, Stoppino G, Panella C. Infliximab single administration followed by acute liver injury. Inflamm Bowel Dis 2006; 12: 1089-91. (28 year old man with ulcerative colitis developed jaundice 9 days after initial infusion of infliximab [peak bilirubin ~6.5 mg/dL, ALT 4 times ULN], resolving within 6 weeks). 17075352
Ierardi E, Della Valle N, Nacchiero MC, De Francesco V, Stoppino G, Panella C. Onset of liver damage after a single administration of infliximab in a patient with refractory ulcerative colitis. Clin Drug Investig 2006; 26: 673-6. (Authors report same case as described in Inflamm Bowel Dis 2006). 17163303
Millonig G, Kern M, Ludwiczek O, Nachbaur K, Vogel W. Subfulminant hepatitis B after infliximab in Crohn's disease: need for HBV-screening? World J Gastroenterol 2006; 12: 974-6. (50 year old man with Crohn disease developed acute hepatitis 1 month after 3rd infusion of infliximab [bilirubin 2.2 rising to 35 mg/dL, ALT 983 U/L, GGT 109 U/L] found to have HBsAg, IgM anti-HBc, anti-HBe and high levels of HBV DNA, improved rapidly on lamivudine therapy and stopping infliximab; testing of stored serum collected before therapy showed that he was HBsAg positive). 16521231
Roux CH, Brocq O, Breuil V, Albert C, Euller-Ziegler L. Safety of anti-TNF-alpha therapy in rheumatoid arthritis and spondyloarthropathies with concurrent B or C chronic hepatitis. Rheumatology (Oxford) 2006; 45: 1294-7. (Retrospective analysis of 6 patients with chronic hepatitis and inflammatory arthritis treated with anti-TNF agents for 3-39 months, none had risen in ALT or viral levels during therapy, but 3 with hepatitis B were also on lamivudine). 16603583
Sánchez Carazo JL, Mahiques Santos L, Oliver Martinez V. Safety of etanercept in psoriasis: a critical review. Drug Saf 2006; 29: 675-85. (Review of safety of etanercept focusing upon psoriasis; no discussion of hepatotoxicity). 16872241
Soto-Fernández S, González-Carro P, De Pedro-Esteban A, Legaz-Huidobro ML, Pérez-Roldán F, Roncero Garcia-Escribano O, Valbuena-González M, et al. [Infliximab-induced hepatitis in a patient with Crohn's disease]. Gastroenterol Hepatol 2006; 29: 321-2. Spanish. PMID: 16733041 (43 year old woman with Crohn disease developed asymptomatic elevations in ALT [289 U/L] after third infusion of infliximab, resolving rapidly, but more severe recurrence and symptoms upon restarting infusions 6 months later [ALT 1497 U/L, Alk P 71 U/L, bilirubin 0.6 mg/dL], resolving within a few months; all viral and autoimmune markers were negative).
Wahie S, Alexandroff A, Reynolds NJ. Hepatitis: a rare, but important, complication of infliximab therapy for psoriasis. Clin Exp Dermatol 2006; 31: 460-1. (64 year old man with psoriasis developed enzyme elevations [ALT 569 U/L, GGT 77 U/L, bilirubin normal] 1 week after a second infusion of infliximab, which resolved within 4 weeks and did not recur with etanercept therapy). 16681606
Nathan DM, Angus PW, Gibson PR. Hepatitis B and C virus infections and anti-tumor necrosis factor-. therapy: guidelines for clinical approach. J Gastro Hepatol 2006; 31: 1366-71. (Review and proposed guidelines for use of anti-TNF therapy in patients with underlying chronic viral hepatitis; recommended screening for HBV and HCV, careful monitoring during therapy and prophylaxis or early intervention with lamivudine in HBsAg-positive patients). 16911678
Rokhsar C, Rabhan N, Cohen SR. Etanercept monotherapy for a patient with psoriasis, psoriatic arthritis, and concomitant hepatitis C infection. J Am Acad Dermatol 2006; 54: 361-2. (53 year old man with severe psoriasis and hepatic fibrosis caused by methotrexate and hepatitis C responded well to etanercept, while HCV RNA levels were unchanged). 16443079
Cecchi R, Bartoli L. Psoriasis and hepatitis C treated with anti-TNF alpha therapy (etanercept). Dermatol Online J 2006; 12: 4. (45 year old man with psoriasis and hepatitis C was treated with etanercept for 12 months and had no change in serum enzyme or HCV RNA levels). 17459290
De Simone C, Paradisi A, Capizzi R, Carbone A, Siciliano M, Amerio PL. Etanercept therapy in two patients with psoriasis and concomitant hepatitis C. J Am Acad Dermatol 2006; 54: 1102-4. (Letter in response to Magliocco [2004] reporting two patients with psoriasis and hepatitis C who tolerated 12 months of etanercept therapy, with no change in serum tests and slight decrease in HCV RNA levels). 16713482
Calabrese LH, Zein NN, Vassilopoulos D. Hepatitis B virus(HBV) reactivation with immunosuppressive therapy in rheumatic diseases: assessment and preventive strategies. Ann Rheum Dis 2006; 65: 983-9. (Review of the problem of reactivation of hepatitis B in patients with rheumatic diseases treated with immunosuppressive agents, with recommendations on prevention). 16627542
Koike R, Takeuchi T, Eguchi K, Miyasaka N; Japan College of Rheumatology. Update on the Japanese guidelines for the use of infliximab and etanercept in rheumatoid arthritis. Mod Rheumatol 2007; 17: 451-8. (Review of guidelines for the use of infliximab and etanercept in rheumatoid arthritis; no mention of hepatotoxicity or need to screen for hepatitis B). 18084695
Vassilopoulos D, Calabrese LH. Risks of immunosuppressive therapies including biologic agents in patients with rheumatic diseases and co-existing chronic viral infections. Curr Opin Rheumatol 2007; 19: 619-25. (Review of use of anti-TNF agents in patients with chronic hepatitis B, C and HIV infection). 17917544
Sakellariou GT, Chatzigiannis I. Long-term anti-TNFalpha therapy for ankylosing spondylitis in two patients with chronic HBV infection. Clin Rheumatol 2007; 26: 950-2. (Two patients with ankylosing spondylitis and inactive HBsAg carrier state who were treated with infliximab; 43 year old man developed reactivation after 14 weeks [ALT 49 U/L, HBV DNA positive] and was successfully treated with lamivudine; 41 year old man had ALT elevations [85 U/L], but no reactivation even when later switched to etanercept). 16865308
García Aparicio AM, Rey JR, Sanz AH, Alvarez JS. Successful treatment with etanercept in a patient with hepatotoxicity closely related to infliximab. Clin Rheumatol 2007; 26: 811-3. (48 year old man with ankylosing spondylitis developed mild ALT elevations [60 U/L] after second and higher levels [ALT 382 rising to 656 U/L, Alk P 166 U/L, bilirubin 0.6 mg/dL, ANA negative] after third and fourth infusion of infliximab, with no recurrence on switching to etanercept: Case 2). 16550301
Hansen RA, Gartlehner G, Powell GE, Sandler RS. Serious adverse events with infliximab: analysis of spontaneously reported adverse events. Clin Gastroenterol Hepatol 2007; 5: 729-35. (Analysis of 15,763 spontaneous, postmarketing adverse event reports attributed to infliximab found that reports of lymphoma and serious infections were more common than could be expected; no mention of rates of reporting liver injury, jaundice or hepatitis). 17481964
Linardaki G, Katsarou O, Ioannidou P, Karafoulidou A, Boki K. Effective etanercept treatment for psoriatic arthritis complicating concomitant human immunodeficiency virus and hepatitis C virus infection. J Rheumatol 2007; 34: 1353-5. (45 year old man with HIV-HCV coinfection and psoriasis was successfully treated with etanercept without worsening of hepatitis while on antiretroviral therapy; ALT levels remained normal, but serial HCV RNA levels were not provided). 17552060
Madonia S, Orlando A, Scimeca D, Olivo M, Rossi F, Cottone M. Occult hepatitis B and infliximab-induced HBV reactivation. Inflamm Bowel Dis 2007; 13: 508-9. (41 year old woman developed acute hepatitis with HBsAg, anti-HBe and HBV DNA after restarting infliximab and prednisone [25 mg/day] for Crohn disease [peak bilirubin 5.5 mg/dL, ALT 10 times ULN], resolving within 2 months with clearance of HBsAg; was known to have been HBsAg negative, but authors suspected HBV reactivation and reverse seroconversion, although anti-HBc and anti-HBs status before therapy was not known). 17206687
Sandborn WJ, Feagan BG, Stoinov S, Honiball PJ, Rutgeerts P, Mason D, Bloomfield R, et al.; PRECISE 1 Study Investigators. Certolizumab pegol for the treatment of Crohn's disease. N Engl J Med 2007; 357: 228-38. (Controlled trial of certolizumab for 26 weeks in 662 adults with Crohn disease; "No clinically significant changes in laboratory values occurred in either study group"; no mention of hepatotoxicity or ALT elevations). 17634458
Ozorio G, McGarity B, Bak H, Jordan AS, Lau H, Marshall C. Autoimmune hepatitis following infliximab therapy for ankylosing spondylitis. Med J Aust 2007; 187: 524-6. (56 year old woman with ankylosing spondylitis developed rising levels of serum enzymes after 3 infusions of infliximab which was stopped after sixth infusion [bilirubin was 5.7 mg/dL, ALT 621 U/L, Alk P 521 U/L, ANA 1:640, SMA 1:2560: all previously negative or normal]; biopsy suggested autoimmune hepatitis, patient improved with prednisolone and stopping infliximab; no follow up beyond 3 months). 17979620
Tobon GJ, Cañas C, Jaller JJ, Restrepo JC, Anaya JM. Serious liver disease induced by infliximab. Clin Rheumatol 2007; 26: 578-81. (Two case reports; 39 and 54 year old women with rheumatoid arthritis developed symptoms after 8 and 17 months of infliximab therapy [bilirubin 15.2 mg/dL and not given, ALT 2560 and 291 U/L, Alk P 840 U/L and not given, ANA 1:640 and 1:160], both were treated with corticosteroids, the first required liver transplant and the second recovered). 16547695
Colbert C, Chavarria A, Berkelhammer C. Fulminant hepatic failure in chronic hepatitis B on withdrawal of corticosteroids. Azathioprine and infliximab for Crohn's disease. Inflamm Bowel Dis 2007; 13: 1453-4. (54 year old man with chronic hepatitis B and Crohn disease developed decompensated cirrhosis while on infliximab and azathioprine; stopping therapy and starting lamivudine was followed by a fatal flare of disease and acute liver failure). 17600380
Marotte H, Fontanges E, Bailly F, Zoulim F, Trepo C, Miossec P. Etanercept treatment for three months is safe in patients with rheumatological manifestations associated with hepatitis C virus. Rheumatology (Oxford) 2007; 46: 97-9. (Among 9 patients with chronic hepatitis C and rheumatologic symptoms treated with etanercept for 3 months, serum ALT levels were stable and HCV RNA levels [present in 5] did not change). 16720634
Aslanidis S, Vassiliadis T, Pyrpasopoulou A, Douloumpakas I, Zamboulis C. Inhibition of TNF alpha does not induce viral reactivation in patients with chronic hepatitis C infection: two cases. Clin Rheumatol 2007; 26: 261-4. (Two patients, 41 year old man and 47 year old woman with chronic hepatitis C were treated with infliximab for 6 and 13 months and had no change in serum ALT, AST or HCV RNA levels [1 had anti-HCV without HCV RNA before therapy]). 16924392
Moum B, Konopski Z, Tufteland KF, Jahnsen J. Occurrence of hepatoxicity and elevated liver enzymes in a Crohn's disease patient treated with infliximab. Inflamm Bowel Dis 2007; 13: 1584-6. (45 year old woman with Crohn disease developed elevations in ALT 5 weeks after starting infliximab [peak bilirubin 3.0 mg/dL, ALT 13 times ULN, Alk P not given, ANA negative], resolving within 6 weeks of stopping). 17663423
Cansu DU, Kalifoglu T, Korkmaz C. Short-term course of chronic hepatitis B and C under treatment with etanercept associated with different disease modifying antirheumatic drugs without antiviral prophylaxis. J Rheumatol 2008; 35: 421-4. (Five patients with inflammatory arthritis, 3 with HCV, 1 with HBV and 1 with both, were treated with etanercept for 12-23 months; none had change in serum ALT or AST levels; viral levels fluctuated, but without a specific pattern). 18203328
Thiéfen G, Morelet A, Heurgué A, Diebold MD, Eschard JP. Infliximab-induced hepatitis: absence of cross-toxicity with etanercept. Joint Bone Spine 2008; 75: 737-9. (48 year old man with ankylosing spondylitis developed rising ALT levels [188 to 393 to 412 U/L] and ANA [1:200 to 1:1600] after 6 infusions of infliximab, which fell to normal 3 months after stopping, and patient was then treated with etanercept for 30 months without changes in ALT levels). 18693125
Dominique L. Liver toxicity of TNF-α antagonists. Joint Bone Spine 2008; 75: 636-8. (Editorial in response to Thiefin [2008]). 18952478
Farah M, Al Rashidi A, Owen DA, Yoshida EM, Reid GD. Granulomatous hepatitis associated with etanercept therapy. J Rheumatol 2008; 35: 349-51. (17 year old woman with an inflammatory arthritis developed abnormal liver tests without symptoms 4 months after restarting etanercept [bilirubin normal, ALT 162 U/L, Alk P 267 U/L], a biopsy showing granulomas and bile duct injury, the injury improving but not resolving completely on stopping etanercept and using ursodiol). 18260163
Fathalla BM, Goldsmith DP, Pascasio JM, Baldridge A. Development of autoimmune hepatitis in a child with systemic-onset juvenile idiopathic arthritis during therapy with etanercept. J Clin Rheumatol 2008; 14: 297-8. (9 year old girl with juvenile idiopathic (rheumatoid) arthritis developed abdominal pain and jaundice 10 months after starting etanercept [bilirubin 12.0 mg/dL, ALT 354 U/L, GGT 388 U/L, ANA 1:640, IgG 3637 mg/dL], stopping etanercept and starting prednisone and azathioprine led to resolution, normal liver tests and negative ANA: Case 1, etanercept). 18824922
Ferri C, Ferraccioli G, Ferrari D, Galeazzi M, Lapadula G, Montecucco C, Triolo G, et al; GISEA Group. Safety of anti-tumor necrosis factor-alpha therapy in patients with rheumatoid arthritis and chronic hepatitis C virus infection. J Rheumatol 2008; 35: 1944-9. (Prospective study in 31 patients with rheumatoid arthritis and hepatitis C treated with anti-TNF agents for 7-44 months [adalimumab 3, etanercept 17; infliximab 11]; mean levels of HCV RNA and ALT did not change; fluctuations occurred in a few patients, but no correlation found between changes in viral RNA and ALT levels). 18688917
García-Simón S, Saliente Callén S, López Avila A, Rabell Iñigo S. [Hepatic cytolysis from infliximab]. Farm Hosp 2008; 32: 250-2. Spanish. PMID: 19128733 (32 year old man with psoriasis developed marked but asymptomatic elevations in serum enzymes after third infusion of infliximab [ALT 1,150 U/L, GGT 185 U/L without change in ANA titer], which resolved 5 months after stopping).
Harada K, Akai Y, Koyama S, Ikenaka Y, Saito Y. A case of autoimmune hepatitis exacerbated by the administration of etanercept in the patient with rheumatoid arthritis. Clin Rheumatol 2008; 27: 1063-6. (50 year old woman with rheumatoid arthritis developed abdominal pain 2 weeks after a first injection of etanercept [bilirubin 1.2 mg/dL, ALT 300 U/L, Alk P 488 U/L, ANA 1:1280]; biopsy suggested autoimmune hepatitis and patient responded to prednisone therapy; may have had mild autoimmune hepatitis before starting therapy and also received diclofenac). 18563514
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, etanercept was implicated in 3 cases, but infliximab was not linked to any). 18955056
Becker H, Willeke P, Domschke W, Gaubitz M. Etanercept tolerance in a patient with previous infliximab-induced hepatitis. Clin Rheumatol 2008; 27: 1597-8. (Letter in response to Harada [2008]; 41 year old woman with seronegative rheumatoid arthritis developed elevated enzymes [ALT 1061 U/L, Alk P 244 U/L] after 3 years of infliximab therapy [ANA rising from 1:160 to 1:640], responding to stopping infliximab and prednisone therapy, later tolerating etanercept without ALT elevations and ANA levels falling to baseline). 18795397
Leak AM, Rincon-Aznar B. Hepatotoxicity associated with etanercept in psoriatic arthritis. J Rheumatol 2008; 35: 2286-7. (50 year old woman with psoriatic arthritis developed jaundice after 2 months of etanercept [50 mg/week] [bilirubin 2.4 mg/dL, ALT ~550 U/L, Alk P ~325 U/L], resolving within 3 months of stopping; but the patient later tolerated a lower dose of etanercept without recurrence of hepatitis, but she continued to have borderline high Alk P levels). 19004062
Marques M, Magro F, Cardoso H, Carneiro F, Portugal R, Lopes J, Costa Santos C. Infliximab-induced lupus-like syndrome associated with autoimmune hepatitis. Inflamm Bowel Dis 2008; 14: 723-5. (34 year old woman with ulcerative colitis developed symptoms and liver tests abnormalities [ALT 412 U/L, Alk P 152, bilirubin normal, ANA 1:3210, IgG 1840 mg/dL] after fourth infusion of infliximab, biopsy showing changes of autoimmune hepatitis; patient worsened despite stopping infliximab for 5 months, then responded to prednisone). 17929297
Ojiro K, Naganuma M, Ebinuma H, Kunimoto H, Tada S, Ogata H, Iwao Y, et al. Reactivation of hepatitis B in a patient with Crohn's disease treated using infliximab. J Gastroenterol 2008; 43: 397-401. (43 year old woman with Crohn disease and HBsAg developed detectable HBV DNA after fourth infusion of infliximab and flare of hepatitis 6 months later despite therapy with lamivudine, resolving after 3 months; later tolerated infliximab with concurrent lamivudine therapy: Case 3). 18592158
Cansu DU, Kalifoglu T, Korkmaz C. Short-term course of chronic hepatitis B and C under treatment with etanercept associated with different disease modifying antirheumatic drugs without antiviral prophylaxis. J Rheumatol 2008; 35: 421-4. (Among 2 patients with HBsAg who received etanercept therapy for 12 and 13 months, serum HBV DNA levels rose minimally [from undetectable to 514 and 36 copies/mL] and ALT levels did not change; in 4 patients with hepatitis C treated with etanercept for 13-234 months, HCV RNA levels rose in 3, but ALT levels were only minimally elevated [<2 times ULN]). 18203328
Levämpi T, Korpela M, Vuolteenaho K, Moilanen E. Etanercept and adalimumab treatment in patients with rheumatoid arthritis and spondyloarthropathies in clinical practice: adverse events and other reasons leading to discontinuation of the treatment. Rheumatol Int 2008; 28: 261-9. (Among 17 patients with inflammatory arthritidies who stopped anti-TNF therapy because of side effects, none were for hepatotoxicity). 17846778
Collazo MH, González JR, Torres EA. Etanercept therapy for psoriasis in a patient with concomitant hepatitis C and liver transplant. P R Health Sci J 2008; 27: 346-7. (49 year old man with psoriasis underwent liver transplantation for liver cancer due to HCV and alcoholic cirrhosis and was treated with etanercept with excellent clinical results, as shown by decreases in ALT and HCV RNA levels [from 822 to 1.3 million IU/mL). 19069362
Cavazzana I, Ceribelli A, Cattaneo R, Franceschini F. Treatment with etanercept in six patients with chronic hepatitis C infection and systemic autoimmune diseases. Autoimmun Rev 2008; 8: 104-6. (Among 6 patients with inflammatory arthritis and anti-HCV who were treated with etanercept, none had worsening of hepatitis and HCV RNA levels changed minimally [174,770 to 348,218 IU/mL]). 19014870
Domm S, Cinatl J, Mrowietz U. The impact of treatment with tumour necrosis factor-alpha antagonists on the course of chronic viral infections: a review of the literature. Br J Dermatol 2008; 159: 1217-28. (Review of literature on efficacy and safety of TNF antagonists in patients with chronic hepatitis B and C recommends screening and monitoring). 18945310
Cassano N, Vena GA. Etanercept treatment in a hemodialysis patient with severe cyclosporine-resistant psoriasis and hepatitis C virus infection. Int J Dermatol 2008; 47: 980-1. (69 year old man on hemodialysis with severe psoriasis and chronic hepatitis C was treated successfully with etanercept without worsening or change in hepatitis C markers or ALT levels). 18937672
Boetticher NC, Peine CJ, Kwo P, Abrams GA, Patel T, Aqel B, Boardman L, et al. A randomized, double-blinded, placebo-controlled multicenter trial of etanercept in the treatment of alcoholic hepatitis. Gastroenterology 2008; 135: 1953-60. (Controlled trial in 48 patients with moderate-to-severe acute alcoholic hepatitis found a higher 6 month mortality rate with etanercept [58%] than placebo therapy [23%]). 18848937
Takeuchi T, Tatsuki Y, Nogami Y, Ishiguro N, Tanaka Y, Yamanaka H, Kamatani N, et al. Postmarketing surveillance of the safety profile of infliximab in 5000 Japanese patients with rheumatoid arthritis. Ann Rheum Dis 2008; 67: 189-94. (Among 5000 patients treated with infliximab for at least 6 months, 28% developed adverse events [6% serious], including 3.9% with hepatobiliary events [0.04% serious], but no details given). 17644554
Carroll MB, Bond MI. Use of tumor necrosis factor-alpha inhibitors in patients with chronic hepatitis B infection. Semin Arthritis Rheum 2008; 38: 208-17. (73 year old woman with rheumatoid arthritis and chronic hepatitis B with high levels of HBV DNA in serum was treated with etanercept and given lamivudine and later adefovir without sustained effects and later followed on no antiviral therapy with no change in liver histology over a 5 year period). 18221983
Zingarelli S, Airò Frassi M, Bazzani C, Scarsi M, Puoti M. Prophylaxis and therapy of HBV infection in 20 patients treated with disease modifying antirheumatic drugs or with biological agents for rheumatic diseases. Reumatismo 2008; 60: 22-7. (Retrospective analysis of results of treating 20 patients with rheumatic conditions and serum HBsAg using immunosuppressive agents, all tolerating therapy well, and reactivation prevented by prophylactic antiviral therapy). 18432322
Montiel PM, Solis JA, Chirinos JA, a Casis B, Sáhez F, Rodríez S. Hepatitis B virus reactivation during therapy with etanercept in an HBsAg-negative and anti-HBs-positive patient. Liver Int 2008; 28: 718-20. (73 year old man with ankylosing spondylitis, amyloidosis and anti-HBc without HBsAg in serum was treated with etanercept and prednisone and developed symptomatic hepatitis 14 months later [bilirubin 2.0 mg/dL, ALT 65 U/L, GGT 121 U/L] with appearance of HBsAg and HBV DNA [1507 U/mL], resolving on lamivudine and later restarting etanercept while continuing lamivudine without reactivation). 18433400
Conde-Taboada A, Muñoz JP, Muñoz LC, Ló-pez Bran E. Infliximab treatment for severe psoriasis in a patient with active hepatitis B virus infection. J Am Acad Dermatol 2009; 60: 1077-80. (36 year old man with psoriasis and chronic hepatitis B successfully treated with combination of lamivudine and infliximab with fall of ALT levels [from 349 to 39 U/L] and HBV DNA [>110,000 to 1266 copies/mL] after 6 months of treatment, but no further follow up). 19467387
Burmester GR, Mease P, Dijkmans BA, Gordon K, Lovell D, Panaccione R, Perez J, et al. Adalimumab safety and mortality rates from global clinical trials of six immune-mediated inflammatory diseases. Ann Rheum Dis 2009; 68: 1863-9. (Among 19,041 patients treated with adalimumab in 36 clinical trials, serious infections occurred in 1-5 patients per year; no discussion of hepatotoxicity or ALT levels). 19147611
Zingarelli S, Frassi M, Bazzani C, Scarsi M, Puoti M, Airò P. Use of tumor necrosis factor-alpha-blocking agents in hepatitis B virus-positive patients: reports of 3 cases and review of the literature. J Rheumatol 2009; 36: 1188-94. (3 patients with rheumatoid arthritis and HBsAg in serum treated with etanercept, infliximab or adalimumab for up to 3 years; 2 with lamivudine prophylaxis did not develop reactivation, 1 without prophylaxis developed mild reactivation at 6 months and was successfully treated with lamivudine; review of literature found reactivation to occur in 12 of 16 patients not given prophylaxis, but only mild rise in HBV DNA in 1 of 7 on lamivudine). 19447932
Robinson H, Walker-Bone K. Anti-TNF-alpha therapy for rheumatoid arthritis among patients with chronic hepatitis B infection. Rheumatology (Oxford) 2009; 48: 448-50. (63 year old woman with rheumatoid arthritis and inactive hepatitis B treated with various combinations of etanercept, adalimumab, prednisone and methotrexate had no evidence of significant reactivation after 2 years of therapy; on review of literature, authors conclude that prophylaxis is not usually necessary). 19223285
Caramaschi P, Bambara LM, Pieropan S, Tinazzi I, Volpe A, Biasi D. Anti-TNFalpha blockers, autoantibodies and autoimmune diseases. Joint Bone Spine 2009; 76: 333-42. (Review of frequency of appearance of autoantibodies and autoimmune conditions during anti-TNF therapy). 19539516
Carlsen KM, Riis L, Madsen OR. Toxic hepatitis induced by infliximab in a patient with rheumatoid arthritis with no relapse after switching to etanercept. Clin Rheumatol 2009; 28: 1001-3. (38 year old woman with rheumatoid arthritis developed rising ALT levels after 7 infusions of infliximab [ALT 234 U/L, bilirubin normal, ANA negative]; resolving with stopping and no recurrence on switching to etanercept). 19370307
Chung SJ, Kim JK, Park MC, Park YB, Lee SK. Reactivation of hepatitis B viral infection in inactive HBsAg carriers following anti-tumor necrosis factor-alpha therapy. J Rheumatol 2009; 36: 2416-20. (Among 103 patients with rheumatoid arthritis or psoriasis treated with anti-TNF agents for 15-52 weeks, 8 were HBsAg-positive, but only 1 suffered reactivation; after third infusion with rise in ALT at week 14 peaking at 1054 U/L, HBV DNA 3.1 million copies/mL, entecavir therapy resulted in prompt improvements). 19797507
Dufour C, Giacchino R, Ghezzi P, Tonelli R, Ferretti E, Pitto A, Pistoia V, et al. Etanercept as a salvage treatment for refractory aplastic anemia. Pediatr Blood Cancer 2009; 52: 522-5. (17 year old man with aplastic anemia and chronic hepatitis C developed mild, transient ALT elevations [peak 176 U/L] during etanercept therapy). 19061218
Fairhurst DA, Sheehan-Dare R. Autoimmune hepatitis associated with infliximab in a patient with palmoplantar pustular psoriasis. Clin Exp Dermatol 2009; 34: 421-2. (22 year old woman with psoriasis developed rising ALT levels after third infusion of infliximab, peaking at ALT 1663 U/L 55 days after last infusion with rising in ANA [1:40 to 1:640] and a liver biopsy suggestive of autoimmune hepatitis, resolving with prednisone therapy; short follow up and no mention of bilirubin levels). 19309375
Kluger N, Girard C, Guillot B, Bessis D. Efficiency and safety of etanercept after acute hepatitis induced by infliximab for psoriasis. Acta Derm Venereol 2009; 89: 332-4. (46 year old woman with psoriasis developed rise in ALT [369 U/L] after a fourth infusion of infliximab with negative ANA and bilirubin of 1.5 mg/dL, resolving within 6 weeks of stopping and no recurrence with etanercept). 19479148
Li S, Kaur PP, Chan V, Berney S. Use of tumor necrosis factor-alpha(TNF-alpha) antagonists infliximab, etanercept, and adalimumab in patients with concurrent rheumatoid arthritis and hepatitis B or hepatitis C: a retrospective record review of 11 patients. Clin Rheumatol 2009; 28: 787-91. (Retrospective analysis of 11 patients with rheumatoid arthritis and either hepatitis B [n=3] or C [n=8] during 3 to 60 months anti-TNF therapy, 3 had transient minimal ALT elevations [peak levels 51, 73 and 51 U/L] without symptoms or jaundice). 19291350
Massarotti M, Marasini B. Successful treatment with etanercept of a patient with psoriatic arthritis after adalimumab-related hepatotoxicity. Int J Immunopathol Pharmacol 2009; 22: 547-9. (46 year old man with psoriatic arthritis developed rising ALT levels [19 to 96 to 252 U/L] 2 months after starting adalimumab, with resolution within 2 months of stopping and no recurrence after switching to etanercept). 19505409
Murakami A, Tanaka Y, Ueda M, Nagano Y, Kunisaki R, Morimoto M, Enaka M, et al. Hepatocellular carcinoma occurring in a young Crohn's disease patient. Pathol Int 2009; 59: 492-6. (25 year old man with 12 year history of Crohn disease developed hepatocellular carcinoma [HCC] without cirrhosis approximately one year after starting infliximab; no other risk factors identified; review of literature identified 7 cases of HCC in patients with Crohn disease, mean age 20 years, all had received azathioprine and 2 infliximab, none had cirrhosis or viral hepatitis). 19563414
Wetter DA, Davis MD. Lupus-like syndrome attributable to anti-tumor necrosis factor alpha therapy in 14 patients during an 8-year period at Mayo Clinic. Mayo Clin Proc 2009; 84: 979-84. (Retrospective analysis of 14 cases of lupus-like syndrome arising during anti-TNF therapy [13 infliximab, 1 adalimumab] over 8 year period; all were ANA positive and most had anti-dsDNA, onset with rash, serositis, fatigue, arthralgias, oral ulcers, but no renal or CNS involvement, all improved on stopping and tolerated other, but not the same anti-TNF agent; no hepatic manifestations mentioned). 19880688
Rodríguez Gil FJ, Martínez Crespo JJ, García Belmonte D, Nicolás de Prado I, de Prado Serrano R. [Jaundice in a patient treated with etanercept]. Gastroenterol Hepatol 2009; 32: 584-5. Spanish. PMID: 19523718 (62 year old woman with primary biliary cirrhosis on ursodiol with mild elevations in Alk P and bilirubin was started on etanercept for psoriasis and 2 months later developed deepening jaundice despite improvements in Alk P and ALT; bilirubin rose gradually to 12.7 mg/dL 5 months after stopping and subsequently fell to baseline as Alk P and ALT levels rose).
Shao LM, Chen MY, Cai JT. Meta-analysis: the efficacy and safety of certolizumab pegol in Crohn's disease. Aliment Pharmacol Ther 2009; 29: 605-14. (Metaanalysis of safety in 3 controlled trials of certolizumab in 1313 patients with Crohn disease; no increase in serious adverse events except for infections, but no specific data on rates of ALT elevation or liver injury provided). 19183161
Smolen J, Landewé RB, Mease P, Brzezicki J, Mason D, Luijtens K, van Vollenhoven RF, et al. Efficacy and safety of certolizumab pegol plus methotrexate in active rheumatoid arthritis: the RAPID 2 study. A randomised controlled trial. Ann Rheum Dis 2009; 68: 797-804. (Controlled trial of methotrexate with or without certolizumab in 619 patients with rheumatoid arthritis; ALT elevations occurred in 5% of patients on methotrexate alone vs 2% on the combination; 5 cases of tuberculosis on certolizumab, but no mention of clinically apparent liver injury). 19015207
Charpin C, Guis S, Colson P, Borentain P, Mattéi JP, Alcaraz P, Balandraud N, et al. Safety of TNF-blocking agents in rheumatic patients with serology suggesting past hepatitis B state: results from a cohort of 21 patients. Arthritis Res Ther 2009; 11: R179. (21 patients with rheumatic conditions who had anti-HBc without HBsAg in serum and were monitored during 7-56 months of therapy with infliximab [4], etanercept [14] or adalimumab [2]; anti-HBs titers decreased minimally, and no patient developed HBV DNA or HBsAg or features of reactivation). 19941642
Frankel AJ, Van Voorhees AS, Hsu S, Korman NJ, Lebwohl MG, Bebo BF Jr, Gottlieb AB; National Psoriasis Foundation. Treatment of psoriasis in patients with hepatitis C: from the Medical Board of the National Psoriasis Foundation. J Am Acad Dermatol 2009; 61: 1044-55. (Recommend that infliximab and etanercept be considered second line agents in patients with psoriasis and hepatitis C, and conclude that more studies are needed). 19811848
Prignano F, Zanieri F, Milani S, Lotti T. Switch from etanercept to efalizumab in a psoriatic patient with HCV infection: a case report. Dermatol Ther 2009; 22: 386-90. (40 year old man with severe psoriasis and chronic hepatitis C was treated with etanercept and then efalizumab for six months without worsening of hepatitis or significant change in HCV RNA levels). 19580583
Giannitti C, Benucci M, Caporali R, Manganelli S, Bellisai F, Sebastiani GD, Galeazzi M. Efficacy and safety of anti-TNF-alpha therapy combined with cyclosporine A in patients with rheumatoid arthritis and concomitant hepatitis C virus infection. Int J Immunopathol Pharmacol 2009; 22: 543-6. (7 patients with rheumatoid arthritis and chronic hepatitis C were treated with cyclosporine and either etanercept or adalimumab and had clinical improvements with no worsening of liver disease, but instead mild decreases in ALT [38 to 26 U/L] and HCV RNA levels [7.1 to 2.3 million IU/mL]). 19505408
Wendling D, Di Martino V, Prati C, Toussirot E, Herbein G. Spondyloarthropathy and chronic B hepatitis. Effect of anti-TNF therapy. Joint Bone Spine 2009; 76: 308-11. (Four patients with chronic hepatitis B and spondylitis treated with infliximab or etanercept; two who did not receive prophylaxis with lamivudine developed rising HBV DNA levels within a month of starting therapy, which then responded to lamivudine therapy). 19346146
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. Life threatening liver disease during treatment with monoclonal antibodies. BMJ 2009; 338: b508. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF] and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow, but eventual recovery). 19224957
Shale MJ, Seow CH, Coffin CS, Kaplan GG, Panaccione R, Ghosh S. Review article: chronic viral infection in the anti-tumour necrosis factor therapy era in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 20-34. (Extensive review of literature on effects of anti-TNF therapies on underlying chronic hepatitis B and C; among 28 HBV-infected patients, reactivation was common in those not on antiviral therapy, more frequent with monoclonal antibodies than etanercept; among 110 HCV-infected patients, little evidence of worsening of disease and in some instances a decrease in HCV RNA levels). 19681818
Mancini S, Amorotti E, Vecchio S, Ponz de Leon M, Roncucci L. Infliximab-related hepatitis: discussion of a case and review of the literature. Intern Emerg Med 2010 (33 year old man with psoriasis developed fatigue and ALT elevations followed by jaundice after a third infusion of infliximab [bilirubin 3.7 mg/dL, ALT 2132 U/L, Alk P 594 U/L, ANA 1:320 and positive anti-dsDNA], responding to corticosteroids [becoming ANA negative], which were discontinued without relapse). 20107930
Smith LS, Nelson M, Dolder CR. Certolizumab pegol: a TNF-{alpha} antagonist for the treatment of moderate-to-severe Crohn's disease. Ann Pharmacother 2010; 44: 333-42. (Review of structure, mechanism of action, pharmacology, safety and efficacy of certolizumab focusing upon Crohn disease; no mention of liver injury or ALT elevations). 20118143
Lichtenstein GR, Thomsen OØ, Schreiber S, Lawrance IC, Hanauer SB, Bloomfield R, Sandborn WJ; Precise 3 Study Investigators. Continuous therapy with certolizumab pegol maintains remission of patients with Crohn's disease for up to 18 months. Clin Gastroenterol Hepatol 2010; 8: 600-9. (Among 241 patients with Crohn disease continued on certolizumab for up to 80 weeks, 2 patients developed tuberculosis, 1 a lupus-like syndrome, 16 [11%] ANA and 4 [2%] anti-dsDNA reactivity; no mention of liver injury or ALT elevations). 20117244
Sokolove J, Strand V, Greenberg JD, Curtis JR, Kavanaugh A, Kremer JM, Anofrei A, et al.; CORRONA Investigators. Risk of elevated liver enzymes associated with TNF inhibitor utilisation in patients with rheumatoid arthritis. Ann Rheum Dis 2010; 69: 1612-7. (Retrospective analysis of ALT and AST elevations among 6861 patients with rheumatoid arthritis enrolled in a North American database receiving TNF inhibitors followed for an average of 1.5 years with ~1.7 determinations yearly; any elevation of ALT or AST occurred in 5.4% of visits, >2 times ULN in 0.6%, >5 times ULN in 0.1%; rates slightly higher for those on infliximab alone or combined with methotrexate and leflunomide). 20448284
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of the hepatotoxicity of drugs used to treat inflammatory bowel disease focusing upon sulfasalazine, thiopurines, TNF inhibitors, and methotrexate). 20926880
Poulin Y, Thérien G. Drug-induced hepatitis and lupus during infliximab treatment for psoriasis: case report and literature review. J Cutan Med Surg 2010; 14: 100-4. (40 year old woman with psoriasis developed raised ALT after 22 weeks of infliximab treatment [5 infusions], with rise in ALT to 136 and then 536 U/L and symptoms of rash, arthralgias and joint swelling, positive ANA [1:60] and liver biopsy showing chronic hepatitis, resolving with 4 weeks of prednisone therapy and no recurrence in subsequent 4 years). 20338127
Haennig A, Bonnet D, Thebault S, Alric L. Infliximab-induced acute hepatitis during Crohn's disease therapy: absence of cross-toxicity with adalimumab. Gastroenterol Clin Biol 2010; 34: e7-8. (46 year old man with Crohn disease developed elevations in ALT [284 and 528 U/L] without Alk P and bilirubin elevations or symptoms after first 3 doses of infliximab, falling to normal in 3 months and not recurring during 6 months of adalimumab therapy). 20189334
Cravo M, Silva R, Serrano M. Autoimmune hepatitis induced by infliximab in a patient with Crohn's disease with no relapse after switching to adalimumab. BioDrugs 2010; 24 Suppl 1:25-7. (38 year old woman with Crohn disease, was on and off infliximab for 8 years, developed abnormal liver tests [bilirubin normal, ALT 191 U/L, ANA 1:640], responding to prednisolone and azathioprine within 12 weeks and later treated with adalimumab without worsening of liver disease, but on long term azathioprine [50 mg/day]). 21175232
Katsanos KH, Tsianos VE, Zois CD, Zioga H, Vagias I, Zervou E, Christodoulou DK, et al.; Northwest Greece IBD Study Group. Inflammatory bowel disease and hepatitis B and C in Western Balkans: a referral centre study and review of the literature. J Crohns Colitis 2010; 4: 450-65. (Among 482 patients with inflammatory bowel disease, 11 had HBV and 4 HCV, antiviral therapy for which did not worsen the underlying bowel disease). 21122543
Song MS, Lee SB, Sohn S, Oh JH, Yoon KL, Han JW, Kim CH. Infliximab treatment for refractory Kawasaki disease in Korean children. Korean Circ J 2010; 40: 334-8. (Among 16 children with Kawasaki disease treated with infliximab, one 4 month old boy developed an acute hepatitis followed by cholecystitis during therapy). 20664742
Goujon C, Dahel K, Bérd F, Guillot I, Gunera-Saad N, Nicolas JF. Autoimmune hepatitis in two psoriasis patients treated with infliximab. J Am Acad Dermatol 2010; 63: e43-4. (Two cases of autoimmune hepatitis during infliximab therapy, 37 and 51 year old men with psoriasis developed symptoms 4-6 weeks after a third infusion [bilirubin 0.8 and 3.2 mg/dL, ALT 1126 and 768 U/L, Alk P 181 and 391 U/L, ANA 1:200 and 1:2560], one resolving upon stopping and one after treatment with ursodiol, corticosteroids and azathioprine). 20633783
Fotiadou C, Lazaridou E, Ioannides D. Safety of anti-tumour necrosis factor-α agents in psoriasis patients who were chronic hepatitis B carriers: a retrospective report of seven patients and brief review of the literature. J Eur Acad Dermatol Venereol 2011; 25: 471-4. (Seven patients with psoriasis and HBsAg carrier state were treated with adalimumab, etanercept or infliximab for 6-24 months with lamivudine prophylaxis and none suffered reactivation, HBV DNA being undetectable or present at low levels). 20561122
Carroll MB, Forgione MA. Use of tumor necrosis factor alpha inhibitors in hepatitis B surface antigen-positive patients: a literature review and potential mechanisms of action. Clin Rheumatol 2010; 29: 1021-9. (Review of literature on anti-TNF therapy in patients with hepatitis B identified 35 cases, 7 cases of reactivation occurred, including 7 of 17 on infliximab, but none of 12 on etanercept or 6 on adalimumab; 18 received lamivudine, but only 7 as prophylaxis). 20556450
Caporali R, Bobbio-Pallavicini F, Atzeni F, Sakellariou G, Caprioli M, Montecucco C, Sarzi-Puttini P. Safety of tumor necrosis factor alpha blockers in hepatitis B virus occult carriers (hepatitis B surface antigen negative/anti-hepatitis B core antigen positive) with rheumatic diseases. Arthritis Care Res (Hoboken) 2010; 62: 749-54. (Among 732 patients treated with anti-TNF agents, 5 had HBsAg and were given prophylaxis with lamivudine and 67 had anti-HBc without HBsAg [25 on infliximab, 23 etanercept, 19 adalimumab], none of whom developed HBsAg or reactivation during an average follow up of 3.5 years). 20535784
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to infliximab or other anti-TNF agents). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children, included 60 due to infliximab making it rank 18th in frequency). 21039766
Gandhi RK, Pickup T, Sheth PB. Is etanercept safe for treating plaque psoriasis in a patient with chronic hepatitis C virus infection? Arch Dermatol 2010; 146: 1151-2. (58 year old man with severe psoriasis and hepatitis C was treated successfully with etanercept and was reported to become HCV RNA negative during treatment). 20956650
Garavaglia MC, Altomare G. Etanercept therapy in patients with psoriasis and concomitant HCV infection. Int J Immunopathol Pharmacol 2010; 23: 965-9. (5 patients with psoriasis and chronic hepatitis C were treated with etanercept for up to 2 years; HCV RNA and ALT levels changed minimally in 4 and rose in 1 who was then treated with peginterferon and ribavirin). 20943071
Prestinari F, Ferguglia G, Laria G. Etanercept in a patient with severe psoriasis and latent viral hepatic disease and latent tuberculosis. Am J Clin Dermatol 2010; 11 Suppl 1: 57-8. (63 year old man with psoriasis, tuberculin positivity and anti-HBc without HBsAg was treated with isoniazid and etanercept without reactivation or appearance of liver injury). 20586514
Bordas X, Martín Sala S. [Etanercept and chronic infection by HCV and HBV]. Actas Dermosifiliogr. 2010; 101 Suppl 1: 82-7. Spanish. PMID: 20492886 (Review of the safety of antirheumatic agents in patients with chronic viral hepatitis, and case report of 55 year old woman with psoriasis and chronic hepatitis B treated with lamivudine and etanercept with no worsening of liver disease and improvement in psoriasis).
Vassilopoulos D, Apostolopoulou A, Hadziyannis E, Papatheodoridis GV, Manolakopoulos S, Koskinas J, Manesis EK, et al. Long-term safety of anti-TNF treatment in patients with rheumatic diseases and chronic or resolved hepatitis B virus infection. Ann Rheum Dis 2010; 69: 1352-5. (Among 131 patients with rheumatic conditions treated with anti-TNF, 14 had HBsAg [all were given prophylactic anti-HBV therapy], 19 had anti-HBs alone [from vaccination] and 19 anti-HBc [from previous infection]; during an average of 2 years of therapy, one patient with HBsAg on lamivudine developed rising titers of HBV DNA and was successfully treated with tenofovir, while all others had no change in serologic status or ALT levels). 20472596
Paradisi A, Caldarola G, Capizzi R, Siciliano M, Annichiarico E, Vecchio FM, Amerio PL, et al. Safety of etanercept in patients with psoriasis and hepatitis C virus assessed by liver histopathology: preliminary data. J Am Acad Dermatol 2010; 62: 1067-9. (Two men, ages 43 and 62 years, with severe psoriasis and chronic hepatitis C were treated with etanercept; monitoring of serum ALT and HCV RNA levels and liver histology showed no change during 12 months of therapy). 20466184
Kim YJ, Bae SC, Sung YK, Kim TH, Jun JB, Yoo DH, Kim TY, et al. Possible reactivation of potential hepatitis B virus occult infection by tumor necrosis factor-alpha blocker in the treatment of rheumatic diseases. J Rheumatol 2010; 37: 346-50. (Among 266 Korean patients with rheumatic conditions receiving anti-TNF therapy, 8 had HBsAg and 88 anti-HBc without HBsAg; 2 of the 8 HBsAg-positive patients developed reactivation and ALT elevations were more common in the anti-HBc-positive group [16%] than the antibody-negative group [6%], but reactivation was not demonstrated and clinical features were not given). 20008922
Féau S, Causse X, Corondan A, Michenet P, Autret-Leca E. [Acute drug-induced hepatitis during adalimumab and ibuprofen treatment]. Gastroenterol Clin Biol 2010; 34: 420-2. French. PMID: 20494537 (61 year old man with rheumatoid arthritis on adalimumab for 15 months and occasional ibuprofen developed hepatitis [bilirubin 2.9 mg/dL, ALT 2491 U/L, Alk P 292 U/L, ANA negative], resolving within 4 months of stopping medications and increasing prednisone dose)
Adar T, Mizrahi M, Pappo O, Scheiman-Elazary A, Shibolet O. Adalimumab-induced autoimmune hepatitis. J Clin Gastroenterol 2010; 44: e20-2. (36 year old woman with psoriasis and Crohn disease developed nausea after starting adalimumab, and after 3 months liver tests were found to be abnormal [bilirubin 0.7 mg/dL, ALT 1265 U/L, Alk P 102 U/L, ANA 1:80], resolving within 2 months of stopping therapy and starting prednisone and azathioprine). 19593165
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. PubMed Citation (Among 261 cases of autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, 24 were attributed to drugs, 11 to minocycline, 11 to nitrofurantoin, but none due to anti-TNF agents; all responded to corticosteroid therapy and did not relapse when withdrawn). 20512992
Kuroda T, Wada Y, Kobayashi D, Sato H, Murakami S, Nakano M, Narita I. Effect of etanercept and entecavir in a patient with rheumatoid arthritis who is a hepatitis B carrier: a review of the literature. Rheumatol Int 2010 [Epub] PMID: (48 year old woman with rheumatoid arthritis and inactive hepatitis B was treated with entecavir and etanercept with good response and no evidence of reactivation of hepatitis B). 20062998
Ventura F, Gomes J, Duarte Mda L, Fernandes JC, Brito C. Efficacy and safety of etanercept in patients with psoriasis and hepatitis C. Eur J Dermatol 2010; 20: 808-9. (Two patients, a 35 year old man and 47 year old woman with both psoriasis and chronic hepatitis C were treated with etanercept with no change in serum ALT [36 to 44 U/L and 40 to 36 U/L], while HCV RNA levels increased in one and decreased in the other). 20923749
Koike T, Harigai M, Inokuma S, Ishiguro N, Ryu J, Takeuchi T, Tanaka Y, et al. Postmarketing surveillance of safety and effectiveness of etanercept in Japanese patients with rheumatoid arthritis. Mod Rheumatol 2011; 21: 343-51. (Summary of 6 month postmarketing surveillance of 13,894 Japanese patients with rheumatoid arthritis treated with etanercept; adverse events were reported in 31% and were severe in 6.2%, severe reactions including pneumonia and interstitial lung disease; abnormal liver tests were reported in 328 patients [2.4%], which were severe in 15 [0.1%]). 21264488
Stine JG, Bass M, Ibrahim D, Khokhar OS, Lewis JH. Dermatologists' awareness of and screening practices for hepatitis B virus infection before initiating tumor necrosis factor-α inhibitor therapy. South Med J 2011; 104: 781-8. (Results of email questionnaire sent to 1,000 US dermatologists found that 52% of 62 respondents were aware of guidelines for screening for HBV before using anti-TNF agents, but only 42% routinely screened patients and none of the 62 had ever seen a case of HBV reactivation). 22089354
Pérez-Alvarez R, Díaz-Lagares C, García-Hernández F, Lopez-Roses L, Brito-Zerón P, Pérez-de-Lis M, Retamozo S, et al.; BIOGEAS Study Group. Hepatitis B virus (HBV) reactivation in patients receiving tumor necrosis factor (TNF)-targeted therapy: analysis of 257 cases. Medicine (Baltimore) 2011; 90: 359-71. (Systematic review of literature identified 257 patients with preexisting HBV markers who received anti-TNF therapy, reactivation occurred in 39% of 89 patients with HBsAg [5 had acute liver failure and 4 died], but only 5% of 168 with anti-HBc without HBsAg [1 died]; lamivudine prophylaxis decreased, but did not eliminate reactivation [62% vs 23% in HBsAg carriers]). 22033451
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of literature identified 153 patients with chronic hepatitis C treated with anti-TNF agents, mostly etanercept, with only 1 with definite worsening of disease on treatment). 21690185
Doyle A, Forbes G, Kontorinis N. Autoimmune hepatitis during infliximab therapy for Crohn's disease: a case report. J Crohns Colitis 2011; 5: 253-5. (60 year old man with Crohn disease who did not improve on prednisone and azathioprine therapy developed rising levels of ALT 14 weeks after starting infliximab [bilirubin not given, ALT 1307 U/L, Alk P 272 U/L], which resolved on stopping infliximab and starting prednisone). 21575891
Goldfeld DA, Verna EC, Lefkowitch J, Swaminath A. Infliximab-induced autoimmune hepatitis with successful switch to adalimumab in a patient with Crohn's disease: the index case. Dig Dis Sci 2011; 56: 3386-8. (58 year old woman with Crohn disease developed ALT elevations [6 times ULN] 6 months after starting infliximab [peak ALT 210 U/L, ANA 1:2560], resolving within 4 months of stopping and later tolerating adalimumab without recurrence). 21597977
Manzano-Alonso ML, Castellano-Tortajada G. Reactivation of hepatitis B virus infection after cytotoxic chemotherapy or immunosuppressive therapy. World J Gastroenterol 2011; 17: 1531-7. (Review of reactivation of hepatitis B with chemotherapy or immune suppression discusses 11 cases attributed to infliximab and 7 to etanercept). 21472116
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Review of liver injury due to antirheumatic drugs discusses ALT elevations caused by anti-TNF agents and autoimmune hepatitis due to infliximab). 21263458
Doubrawa E, Ricca RA, Malucelli TO, Pizzol VI, Barros DH, Paiva ES. Use of infliximab in a patient with rheumatoid arthritis and chronic hepatitis B. Rev Bras Reumatol 2012; 52: 653-5. (56 year old man with rheumatoid arthritis and HBsAg was treated with infliximab for 15 months while receiving tenofovir and lamivudine for hepatitis B and had no evidence of reactivation). 22885430
Abramson A, Menter A, Perrillo R. Psoriasis, hepatitis B, and the tumor necrosis factor-alpha inhibitory agents: a review and recommendations for management. J Am Acad Dermatol 2012; 67: 1349-61. (Systematic review of the literature on risk of reactivation of hepatitis B in patients with psoriasis on anti-TNF therapy found considerable risk in patients with HBsAg who do not receive antiviral prophylaxis, but no reported cases of reactivation among patients with anti-HBc without HBsAg). 22727462
Titos Arcos JC, Hallal H, Robles M, Andrade RJ. Recurrent hepatotoxicity associated with etanercept and adalimumab but not with infliximab in a patient with rheumatoid arthritis. Rev Esp Enferm Dig 2012; 104: 282-4. (47 year old woman with rheumatoid arthritis was found to have abnormal liver tests 2 years after starting etanercept [ALT 13 times ULN, ANA positive], resolving within 80 days of stopping and recurring 2 months after starting adalimumab [ALT 4 times ULN], but not after switching to infliximab). 22662786
Iwamoto M, Minota S. Successful treatment with very low-dose etanercept in a patient with etanercept-induced liver dysfunction. Rheumatol Int 2011; 31: (37 year old woman with rheumatoid arthritis developed ALT elevations without symptoms 12 weeks after starting etanercept which continued to rise to week 20 [ALT 170 U/L], but later tolerated etanercept at a reduced dose with enzyme elevations). 20349067
Naveau S, Chollet-Martin S, Dharancy S, Mathurin P, Jouet P, Piquet MA, Davion T, et al; Foie-Alcool group of the Association Française pour l'Etude du Foie. A double-blind randomized controlled trial of infliximab associated with prednisolone in acute alcoholic hepatitis. Hepatology 2004; 39: 1390-7. (A prospective randomized controlled trial of infliximab in 36 patients with severe acute alcoholic hepatitis was stopped early because of excess mortality in the infliximab [39%] vs placebo [18%] treated patients, probably due to increased risk of infections). 15122768
Subramaniam K, Chitturi S, Brown M, Pavli P. Infliximab-induced autoimmune hepatitis in Crohn's disease treated with budesonide and mycophenolate. Inflamm Bowel Dis. 2011; 17: E149-50. (33 year old man with Crohn disease developed symptoms and liver test abnormalities 5 months after starting infliximab [bilirubin normal, ALT 1227 U/L, Alk P 132 U/L, ANA 1:1280], resolving only after treatment with budesonide and mycophenolate). 21987301
Viganò M, Degasperi E, Aghemo A, Lampertico P, Colombo M. Anti-TNF drugs in patients with hepatitis B or C virus infection: safety and clinical management. Expert Opin Biol Ther 2012; 12: 193-207. (Systematic review of effects of anti-TNF agents on hepatitis B and C, concluding that patients with hepatitis B should receive antiviral prophylaxis whereas those with hepatitis C need not). 22188392
Grasland A, Sterpu R, Boussoukaya S, Mahe I. Autoimmune hepatitis induced by adalimumab with successful switch to abatacept. Eur J Clin Pharmacol 2012; 68: 895-8. d PMID: 22205272 (35 year old woman with rheumatoid arthritis developed liver enzyme elevations 2 months after switching from etanercept to adalimumab [bilirubin normal, ALT 266 U/L, Alk P normal, ANA 1:80, SMA 1:320], resolving after stopping and increasing dose of prednisone; later tolerating abatacept [anti-CTLA4]).
Di Minno MN, Iervolino S, Peluso R, Russolillo A, Lupoli R, Scarpa R, Di Minno G, et al; CaRRDS Study Group. Hepatic steatosis and disease activity in subjects with psoriatic arthritis receiving tumor necrosis factor-α blockers. J Rheumatol 2012; 39: 1042-6. (48 patients with psoriatic arthritis and hepatic steatosis by ultrasound were monitored prospectively during anti-TNF treatment; steatosis increased in 47% of anti-TNF treated patients, but only 19% of controls). 22422493
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. (Review of hepatotoxicity of antirheumatic agents). 23128910
Kinnunen U, Färkkilä M, Mäkisalo H. A case report: ulcerative colitis, treatment with an antibody against tumor necrosis factor (infliximab), and subsequent liver necrosis. J Crohns Colitis 2012; 6: 724-7. (46 year old woman with ulcerative colitis developed jaundice a month after the second infusion of infliximab [bilirubin 16.6 mg/dL, ALT 1826 U/L, Alk P 283 U/L, INR 3.6, ANA negative], with progressive liver failure and liver transplantation). 22398069
Park SH, Yang SK, Lim YS, Shim JH, Yang DH, Jung KW, et al. Clinical courses of chronic hepatitis B virus infection and inflammatory bowel disease in patients with both diseases. Inflamm Bowel Dis 2012; 18: 2004-10. (Among 4153 Korean patients with inflammatory bowel disease, 134 [3.2%] had HBsAg but only 23 [17%] had abnormal liver tests, but mortality rate was higher in HBsAg-positive than -negative group [5.2% vs 0.4%], with 2 deaths from liver failure and 3 liver cancer). 22337144
Caussé S, Bouquin R, Wylomanski S, Flamant M, Joubert M, Dréno B, Quéreux G. [Infliximab-induced hepatitis during treatment of vulvar Crohn's disease]. Ann Dermatol Venereol 2013; 140: 46-51. French. PMID: 23328360 (29 year old woman with Crohn disease developed ALT elevations 6 days after an initial infusion of infliximab, levels rising to 22 times ULN one month later and remaining elevated until treated with prednisone 2-3 months later).
Efe C. Drug induced autoimmune hepatitis and TNF-α blocking agents: is there a real relationship? Autoimmun Rev 2013; 12: 337-9. (Review of evidence that anti-TNF agents induced autoimmune hepatitis commenting on the rarity of clinically apparent liver injury and the underlying autoimmune diathesis of most treated patients). 22841985
Arai O, Omoto K, Notohara K, Shibata N, Kuboki M, Ikeda H. A case of infliximab-related liver damage -case report and literature review-. Nihon Shokakibyo Gakkai Zasshi 2013; 110: 104-11. (Abstract; 50 year old woman with Behcet disease developed liver injury after the fourth infusion of infliximab, which did not improve despite stopping infliximab, later responding to corticosteroids). 23303236
Lin MV, Blonski W, Buchner AM, Reddy KR, Lichtenstein GR. The influence of anti-TNF therapy on the course of chronic hepatitis C virus infection in patients with inflammatory bowel disease. Dig Dis Sci 2013; 58: 1149-56. (Among 4274 patients with inflammatory bowel disease and 3523 with hepatitis C seen in a single health care system, 37 had both, 5 of whom received anti-TNF, none of whom developed flares of hepatitis C during therapy). 23179145
Weiler-Normann C, Schramm C, Quaas A, Wiegard C, Glaubke C, Pannicke N, Möller S, et al. Infliximab as a rescue treatment in difficult-to-treat autoimmune hepatitis. J Hepatol 2013; 58: 529-34. (11 patients with autoimmune hepatitis that was poorly controlled with conventional medications were treated with infusions of infliximab, with improvements in all and sustained response even after stopping in some; infectious complications were common). 23178709
Navarro R, Vilarrasa E, Herranz P, Puig L, Bordas X, Carrascosa JM, Taberner R, et al. Safety and effectiveness of ustekinumab and antitumour necrosis factor therapy in patients with psoriasis and chronic viral hepatitis B or C: a retrospective, multicentre study in a clinical setting. Br J Dermatol 2013; 168: 609-16. (Among patients with psoriasis and hepatitis B [n=5] or C [n=20], none had significant worsening of disease during courses of ustekinumab [4] or anti-TNF therapy; all patients with hepatitis B received antiviral prophylaxis). 22985451
Kuwabara H, Fukuda A, Tsuda Y, Shibayama Y. Precore mutant hepatitis B virus-associated fulminant hepatitis during infliximab therapy for rheumatoid arthritis. Clin Rheumatol 2013; 32 Suppl 1: S47-9. (73 year old woman with rheumatoid arthritis and HBsAg positivity [HBeAg negative, normal ALT] developed fatal reactivation of hepatitis B after a year of infliximab [bilirubin 15.7 mg/dL, ALT 544 U.L, GGT 130 U/L, HBV DNA and IgM anti-HBc positive], progressing to hepatic failure and death 18 days later). 20379839
Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al; U.S. Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepatol 2013; 11: 558-64. (Description of 6 cases of liver injury attributed to anti-TNF agents [3 infliximab, 2 etanercept, 1 adalimumab] in 5 women and 1 man, mean age 32 years with time to onset of 2 to 52 weeks; 3 were ANA positive and 5 were treated with prednisone; all resolved; review of 28 cases described in the literature, most due to infliximab [26], one resulting in liver transplant). 23333219
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 4 [1 with jaundice] attributed to infliximab [ranking 3rd], for an estimated incidence of 1 per 148 persons exposed). 23419359
Pompili M, Biolato M, Miele L, Grieco A. Tumor necrosis factor-α inhibitors and chronic hepatitis C: a comprehensive literature review. World J Gastroenterol 2013; 19: 7867-73. (Systematic review of the literature on the safety of TNF antagonists in patients with chronic HCV infection identified reports on a total of 216 patients, and only rare instances of worsening of liver disease during therapy). 24307780
Kim E, Bressler B, Schaeffer DF, Yoshida EM. Severe cholestasis due to adalimumab in a Crohn's disease patient. World J Hepatol 2013; 5: 592-5. (39 year old woman with Crohn disease developed jaundice and itching 7 months after adding adalimumab to azathioprine [bilirubin 9.8 mg/dL, ALT 15 U/L, Alk P 183 U/L, ANA negative], biopsy showing bland cholestasis and injury, resolving 10 weeks after stopping both drugs, but later tolerating azathioprine alone). 24179620
Zhang X, Zhang F, Wu D, Bao C, Zhu P, Zhang X, Huang C, et al. Safety of infliximab therapy in rheumatoid arthritis patients with previous exposure to hepatitis B virus. Int J Rheum Dis 2013; 16: 408-12. (Among 234 Chinese patients with rheumatoid arthritis treated with infliximab for 26 weeks, 41 had preexisting antibody to hepatitis B without HBsAg, of whom none developed biochemical or virologic evidence of reactivation during therapy). 23992260
Italian Group for the Study of Inflammatory Bowel Disease, Armuzzi A, Biancone L, Daperno M, Coli A, Pugliese D, Annese V, Aratari A, et al. Adalimumab in active ulcerative colitis: a "real-life" observational study. Dig Liver Dis 2013; 45: 738-43. (Retrospective analysis of the efficacy and safety of adalimumab in ulcerative colitis from 22 Italian centers identified 88 patients; side effects were reported in 12 patents, but none were due to liver injury). 23683530
Colina F, Molero A, Casís B, Martínez-Montiel P. Infliximab-related hepatitis: a case study and literature review. Dig Dis Sci 2013; 58: 3362-7. (52 year old woman with ulcerative colitis developed liver test abnormalities after the 4th infusion of infliximab [bilirubin 0.6 mg/dL, ALT 683 U/L, Alk P 218 U/L, ANA positive], which remained elevated when infliximab was stopped, but became normal with prednisone therapy; discusses 28 cases from 25 publications in the literature). 23645381
Carvalheiro J, Mendes S, Sofia C. Infliximab induced liver injury in Crohn's disease: A challenging diagnosis. J Crohns Colitis 2013 Nov 29. [Epub ahead of print] (24 year old man with Crohn disease developed serum enzyme elevations after a 2nd infusion of infliximab, which increased over the next 5 months [bilirubin not given, peak ALT 211 U/L, Alk P 388 U/L] and then fell back into the normal range 8 months after switching to adalimumab). 24291019
Dang LJ, Lubel JS, Gunatheesan S, Hosking P, Su J. Drug-induced lupus and autoimmune hepatitis secondary to infliximab for psoriasis. Australas J Dermatol 2014 55: 75-9. (47 year old woman with psoriasis had risen in ALT after fourth injection of infliximab [ALT 210 U/L, ANA 1:2560], responding to corticosteroids and later tolerating ustekinumab [anti-IL12 and -IL23]). 23651182
Rossi RE, Parisi I, Despott EJ, Burroughs AK, O'Beirne J, Conte D, Hamilton MI, Murray CD. Anti-tumour necrosis factor agent and liver injury: literature review, recommendations for management. World J Gastroenterol 2014; 20: 17352-9. (Review of the literature on liver injury during anti-TNF therapy stresses that most ALT elevations are mild-to-moderate and self-limiting even with continuation of therapy). 25516646
Olfa H, Aroua G, Wissem M, Wafa BM, Hichem L, Nabil BC, Fethia B, et al. [Fulminant acute hepatitis B after infliximab treatment in Crohn's disease]. Tunis Med 2014; 92: 349-50. French. PMID: 25504398 (23 year old Tunisian man with Crohn disease developed fever and fatigue 5 weeks after the 7th infusion of infliximab [ALT 70 times ULN, bilirubin and Ak P not given, prothrombin index 30%, HBsAg and IgM anti-HBc positive], with progressive liver failure, coma and death within 10 days of presentation; testing before treatment indicated that he was negative for anti-HBc suggesting acute hepatitis B rather than HBV reactivation as the cause).
Yilmaz B, Roach EC, Koklu S. Infliximab leading to autoimmune hepatitis: an increasingly recognized side effect. Dig Dis Sci 2014; 59: 2602-3. (39 year old woman with ankylosing spondylitis developed enzyme elevations after a fourth infusion of infliximab [ALT 500-600 U/L, bilirubin and Alk P not given], responding rapidly to prednisolone and azathioprine therapy; no mention of long term outcome). 25146841
Bonacini M, Ghabril M, Bonkovsky HL. Hepatotoxicity of anti-TNF agents. Dig Dis Sci 2014; 59: 1070-1. (Letter in response to Colina [2013] mentioning results from their 6 cases and literature review [Ghabril 2013]). 24652111
Carvalheiro J, Mendes S, Sofia C. Infliximab induced liver injury in Crohn's disease: a challenging diagnosis. J Crohns Colitis 2014; 8: 436-7. (24 year old man with Crohn disease developed liver enzyme elevations after a second infusion of infliximab [bilirubin not given, ALT 211 U/L, Alk P 388 U/L], biopsy showing chronic hepatitis and cholestasis, improving slowly after switching to adalimumab). 24291019
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; but none were attributed to a TNF antagonist). 24552865
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, et al. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease receiving anti-TNF therapies between 2009 and 2013, 102 developed ALT elevations but half could be attributed to another cause and the 48 attributed to infliximab [45 of 1170: 3%] or adalimumab [3 of 575: 0.5%], 34 patients [71%] recovering despite continuation of therapy, 4 stopping therapy and 10 switching to an alternative agent without suffering recurrence). 25756190
Bauer H, Luxembourger C, Gottenberg JE, Fournier S, Abravanel F, Cantagrel A, Chatelus E, et al.; Club Rhumatismes et Inflammation, a section of the French Society of Rheumatology. Outcome of hepatitis E virus infection in patients with inflammatory arthritidies treated with immunosuppressants: a French retrospective multicenter study. Medicine (Baltimore) 2015; 94: e675. (Survey of French physicians treating patients with rheumatic diseases identified 23 patients who developed acute hepatitis E while being treated with immunosuppressive regimens [10 on anti-TNF, 4 rituximab, 2 abatacept, 2 tocilizumab and 16 receiving methotrexate, 4 leflunomide and 1 cyclosporine]; all recovered and cleared HEV RNA, some after reduction in immunosuppression and 5 with ribavirin therapy). 25860212
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Capkin E, Karkucak M, Cosar AM, Ak E, Karaca A, Gokmen F, Budak BS, Tosun M. Treatment of ankylosing spondylitis with TNF inhibitors does not have adverse effect on results of liver function tests: a longitudinal study. Int J Rheum Dis 2015; 18: 548-52. (Among 94 patients with ankylosing spondylitis treated with infliximab [n=28], adalimumab [n=32] or etanercept [n=34], there was no change in mean ALT levels after 3 and 6 months of therapy). 24612551
Petríková J, Jarčuška P, Svajdler M, Pella D, Macejová Z. Autoimmune hepatitis triggered by adalimumab and allergic reactions after various anti-TNFα therapy agents in a patient with rheumatoid arthritis. Isr Med Assoc J 2015; 17: 256-8. (33 year old woman with rheumatoid arthritis developed fatigue after 3 doses of adalimumab [bilirubin not given, ALT 888 U/L, Alk P 348 U/L, ANA positive], biopsy showing interface hepatitis, resolving with prednisolone; later having allergic reactions to etanercept and certolizumab, but responding to anakinra). 26040057
Shelton E, Chaudrey K, Sauk J, Khalili H, Masia R, Nguyen DD, Yajnik V, Ananthakrishnan AN. New onset idiosyncratic liver enzyme elevations with biological therapy in inflammatory bowel disease. Aliment Pharmacol Ther 2015; 41: 972-9. (Among 1753 patients with inflammatory bowel disease treated with anti-TNF agents, 102 [6%] developed ALT elevations, but half could be attributed to other causes; among 48 with suspected anti-TNF injury [45 infliximab, 3 adalimumab], 34 resolved spontaneously and were able to continue therapy, 10 switched to another agent without recurrence, 4 were treated with corticosteroids). 25756190
Cetkovska P, Lomicova I, Mukensnabl P, Kroes AC. Anti-tumour necrosis factor treatment of severe psoriasis complicated by Epstein-Barr Virus hepatitis and subsequently by chronic hepatitis. Dermatol Ther 2015; 28: 369-72. (38 year old woman with ulcerative colitis developed liver injury after 5th dose of infliximab [bilirubin 20.6 mg/dL, ALT 600 U/L, Alk P 180 U/L, ANA positive, EBV viremia], resolving with galganciclovir therapy, later tolerating adalimumab). 26278774
Rodrigues S, Lopes S, Magro F, Cardoso H, Horta e Vale AM, Marques M, Mariz E, et al. Autoimmune hepatitis and anti-tumor necrosis factor alpha therapy: A single center report of 8 cases. World J Gastroenterol 2015; 21: 7584-8. (Among more than 600 patients treated with anti-TNF agents over a 7 year period, 8 developed autoimmune hepatitis [7 on infliximab, 1 adalimumab]; 3 men, 5 women, most with ANA, 2 symptomatic, no mention of jaundice; all responding to corticosteroids, 2 requiring long term therapy). 26140007
Parra RS, Feitosa MR, Machado VF, Ramalho LN, da Rocha JJ, Feres O. Infliximab-associated fulminant hepatic failure in ulcerative colitis: a case report. J Med Case Rep 2015; 9: 249. (38 year old with ulcerative colitis developed liver injury after 5 doses of infliximab [ALT 408 U/L] with progression to liver failure requiring liver transplantation [bilirubin 23.4 mg/dL, ALT 2177 U/L, Alk P not given, INR 4.1], no mention of ANA or corticosteroid therapy). 26518665
Björnsson ES, Gunnarsson BI, Gröndal G, Jonasson JG, Einarsdottir R, Ludviksson BR, Gudbjörnsson B, Olafsson S. Risk of drug-induced liver injury from tumor necrosis factor antagonists. Clin Gastroenterol Hepatol 2015; 13: 602-8. (Among 11 cases of liver injury from anti-TNF agents identified over a 5 year period in Iceland, 9 were due to infliximab [among 1076 patients treated=1:120], 1 adalimumab [270 treated] and 1 etanercept [430 treated]; 8 women, 3 men; latency 1 to 6 months; 5 were jaundiced [peak bilirubin 0.6-7.6 mg/dL, ALT 169-1658 U/L, Alk P 71-916 U/L], 8 hepatocellular, 2 cholestatic and 1 mixed injury; 8 had ANA, 5 were treated with corticosteroids [only 1 long term], 8 were switched to another anti-TNF agent without recurrence). 25131534
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases [0.7%] were attributed to a tumor necrosis factor antagonist, including 3 to infliximab, 2 etanercept and 1 adalimumab, but none to certolizumab or golimumab). 25754159
Cheng FK, Bridges EE, Betteridge JD. Drug-induced liver injury from initial dose of infliximab. Mil Med 2015; 180: e723-4. (27 year old man with ulcerative colitis developed ALT elevations within days of first infusion of infliximab [ALT 213 U/L, bilirubin and Alk P not given], with rapid resolution and recurrence within days of a second infusion [ALT 474 U/L]). 26032391
Mostamand S, Schroeder S, Schenkein J, Miloh T. Infliximab associated immunomediated hepatitis in children with inflammatory bowel disease. J Pediatr Gastroenterol Nutr 2016 Jan 29. [Epub ahead of print] (2 children, boy age 12 and girl age 15 with ulcerative colitis developed liver test abnormalities 4 to 5 months after starting infliximab [bilirubin 0.5 and not given, ALT 234 and 260 U/L, GGT not given and 117 U/L, both ANA negative], liver biopsies showing inflammation and necrosis, resolving within 1 to 3 months of stopping infliximab). 26835903
Chiu YM, Tang CH, Hung ST, Yang YW, Fang CH, Lin HY. A real-world risk analysis of biological treatment (adalimumab and etanercept) in a country with a high prevalence of tuberculosis and chronic liver disease: a nationwide population-based study. Scand J Rheumatol 2017:46:236-40. 27766916 (Nationwide population-based data on use of adalimumab [n=4049] and etanercept [n=5117] between 2007 and 2011, identified higher rates of serious hepatic events for adalimumab vs etanercept [0.75 vs 0.39 per 100 person years] as well as higher rates of tuberculosis [1.62 vs 0.57 per 100 person-years]).
Parisi I, O'Beirne J, Rossi RE, Tsochatzis E, Manousou P, Theocharidou E, et al. Elevated liver enzymes in inflammatory bowel disease: the role and safety of infliximab. Eur J Gastroenterol Hepatol 2016; 28: 786-91. (In a retrospective analysis of liver test abnormalities in 305 patients with inflammatory bowel disease followed between 2008 and 2013, ALT elevations arose in 36% of patients, only slightly more commonly in those on infliximab [n=176: 39%] than on other agents [n=129: 33%], most elevations being mild and resolving spontaneously). 27015138
Forker R, Escher M, Stange EF. Colitis ulcerosa und fulminantes Leberversagen bei einer 20‑jährigen Patientin [A 20-year-old woman with ulcerative colitis and acute liver failure]. Internist (Berl). 2017;58:982-989. German. PMID: 28271269 (20 year old woman with refractory ulcerative colitis developed fatigue and marked serum enzyme elevations 4 days after an initial infusion of infliximab [bilirubin 1.8 mg/dL, ALT 2685 U/L, GGT 222 U/L, INR 11.0] which fell rapidly with supportive therapy).
Koller T, Galambosova M, Filakovska S, Kubincova M, Hlavaty T, Toth J, Krajcovicova A, et al. Drug-induced liver injury in inflammatory bowel disease: 1-year prospective observational study. World J Gastroenterol. 2017;23:4102-4111. (Among 251 patients with inflammatory bowel disease enrolled in a prospective study with liver test monitoring every 3 months, 66 [22%] had ALT elevations that were usually transient and mild, most commonly in those on infliximab, only 16 patients had ALT elevations above twice normal, only 4 of which persisted, none with symptoms or bilirubin elevations, and all with other possible causes such as alcohol use or obesity). 28652663
Ricciuto A, Kamath BM, Walters TD, Frost K, Carman N, Church PC, Ling SC, et al. New onset autoimmune hepatitis during anti-tumor necrosis factor-alpha treatment in children. J Pediatr. 2018;194:128-135.e1. (17 year old girl with Crohn disease developed abdominal pain 23 weeks [6 infusions] after starting infliximab [bilirubin not given, ALT 359 U/L, GGT 45 U/L, ALT 1:640] resolving after stopping; and review of 659 children treated for inflammatory bowel disease with infliximab at their institution between 2000 and 2015, found ALT elevations in 8% but none developed jaundice or clinically apparent liver injury or required drug discontinuation for liver injury). 29274889
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab induced liver injury, 3 women, 1 man, ages 34 to 59 years, with latency of 1 to 12 months, with hepatocellular pattern of enzyme elevations, 3 with ANA positivity resulting in liver transplant in 3 and death in one). 29564668
Shah P, Larson B, Wishingrad M, Nissen N, Björnsson E, Sundaram V. Now you see it, now you do not: a case of infliximab-induced vanishing bile duct syndrome. ACG Case Rep J. 2019;6:e00134. (63 year old African American man with ulcerative colitis developed jaundice 3 months after starting infliximab [bilirubin 16.0 mg/dL, ALT 1,164 U/L, Alk P 464 U/L] with progressive jaundice despite stopping [peak bilirubin 55.3 mg/dL] and biopsy showing vanishing bile duct syndrome, and requiring liver transplantation 5 weeks after onset). 31620531
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
Bruno CD, Fremd B, Church RJ, Daly AK, Aithal GP, Björnsson ES, Larrey D, et al. HLA associations with infliximab-induced liver injury. Pharmacogenomics J. 2020;20:681-686. (Amng 16 European patients with infliximab-induced liver injury compared to 60 matched controls, genome-wide association studies showed no apparent gene differences but imputation of HLA alleles found a higher carrier rate of B*39:01 in cases [n=4, carrier rate 25%] vs controls [none, estimated 2%). 32024945
Worland T, Chin KL, van Langenberg D, Garg M, Nicoll A. Retrospective study of idiosyncratic drug-induced liver injury from infliximab in an inflammatory bowel disease cohort: the IDLE study. Ann Gastroenterol. 2020;33:162-169. (Among 175 patients with inflammatory bowel disease treated with infliximab at a single Australian referral center, 57 developed ALT elevations, 11 were “possibly” liver injury, one was highly probable - a 60 year old man who developed ALT elevations [298 U/L] after 3 months of treatment that continued for 3 more months [ALT peak 546 U/L, bilirubin normal], falling to normal 13 weeks after stopping infliximab infusions). 32127737
Almeida DE, Costa E, Neves JS, Cerqueira M, Ribeiro AR. Cutaneous vasculitis and granulomatous hepatitis as paradoxical adverse events of Infliximab. Acta Reumatol Port. 2020;45:156-157. English. PMID: 32895360 (58 year old man with psoriatic arthritis developed rash 13 months after starting infliximab accompanied by liver test abnormalities [bilirubin normal, ALT 125 U/L, GGT 512 U/L, Alk P 548 U/L, ANA 1:320] biopsy showing granulomatous hepatitis and skin showing vasculitis, both resolving with stopping therapy and corticosteroid therapy ).
Sagami S, Nishikawa K, Yamada F, Suzuki Y, Watanabe M, Hibi T. Post-marketing analysis for biosimilar CT-P13 in inflammatory bowel disease compared with external data of originator infliximab in Japan. J Gastroenterol Hepatol. 2021;36:2091-2100. (Post-marketing surveillance of 563 Japanese patients treated with an anti-TNF “biosimilar” called CT-P13 and comparison to 396 patients receiving infliximab showed similar rates of liver test abnormalities [18.5% vs 15.4%], most abnormalities resolving without discontinuation). 33450057
Mustafa Alikhan M, Mansoor E, Satyavada S, Greer K, Xin W, Cohen S, Cooper G, et al. Infliximab-induced acute liver failure in a patient with Crohn's disease requiring orthotopic liver transplantation. ACG Case Rep J. 2021;8:e00586. (25 year old man with Crohn disease developed anorexia followed by pruritus and jaundice 2 to 3 months after starting infliximab [bilirubin 10.7 mg/dL, ALT 499 U/L, AST 2776 U/L, ANA 1:80, INR 1.6] biopsy showing acute hepatitis and extensive necrosis and worsened despite methylprednisolone therapy, undergoing liver transplant). 34007859
Jenkins A, Austin A, Hughes K, Sadowski B, Torres D. Infliximab-induced autoimmune hepatitis. BMJ Case Rep. 2021;14:e239944. (31 year old man with refractory ulcerative colitis had a clinical response to infliximab but after 3 months developed elevated liver tests [ALT 130 U/L, bilirubin and Alk P normal, ANA negative] with persistence of ALT elevations [peak 440 U/L] despite stopping therapy, but which rapidly became normal with corticosteroid therapy). 34031069
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enzymes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, mostly with rheumatologic diseases, latency to onset median of 110 days, usually with moderate hepatocellular enzyme elevations and minimal increases in Alk P and bilirubin, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists; one case presented with a cholestatic enzymes that persisted and biopsy showed paucity of bile ducts). 34487751
Meunier L, Malezieux E, Bozon A, Meszaros M, Larrey D. Can azathioprine prevent infliximab-induced liver injury? J Hepatol. 2022;77:553-555. (Letter in response to Bjornsson [2021]: Among 320 patients with inflammatory bowel disease receiving infliximab, two [0.7%] developed hepatitis, both women, ages 40 and 52 years, on infliximab without azathioprine for 4 to 5 months, initial ALT 320 and 318 U/L, with autoimmune features and persistent enzyme elevations despite stopping, with favorable response to corticosteroids; the authors hypothesize that concurrent azathioprine therapy might prevent the immune-mediated hepatitis). 35218814
Núñez F P, Quera R, Bay C, Castro F, Mezzano G. Drug-induced liver injury used in the treatment of inflammatory bowel disease. J Crohns Colitis. 2022;16:1168-1176. (Review of the hepatic adverse events that occur with therapies of inflammatory bowel disease such as sulfasalazine, thiopurines, methotrexate, TNF antagonists, newer monoclonal and small molecule inhibitors, and sphingosine-1-phosphate modulators). 35044449
Eiswerth MJ, Heckroth MA, Ismail A, Gondim DD, Kaufman R. Infliximab-induced vanishing bile duct syndrome. Cureus. 2022;14:e21940. (51 year old man with melanoma developed jaundice 6 weeks after starting infliximab given for pembrolizumab-induced immune colitis [bilirubin 16.1 mg/dL, ALT 1408 U/L, Alk P 579 U/L, INR 1.0], bilirubin rising to 23.0, and liver biopsy showing cholestasis and ductopenia indicative of vanishing bile duct syndrome, treated with corticosteroids with little response). 35273881
Zachou M, Pikramenos K, Panoutsakou M, Lalla E, Androutsakos T. Infliximab (IFX)-biosimilar induced drug-induced liver injury (DILI): a case report. Cureus. 2022;14:e32525. (42 year old woman with Crohn disease started CT-P13 [infliximab biosimilar] after failure of adalimumab and developed abnormal liver tests after 2 infusions [bilirubin 0.5 mg/dL, ALT 234 U/L, Alk P 43 U/L] that resolved with stopping and recurred with restarting [ALT 156 U/L] and she later had a clinical resolve without liver injury to natalizumab). 36654618
Kashima S, Sawada K, Moriichi K, Fujiya M. A case report of drug-induced liver injury due to the infliximab biosimilar CT-P13 on switching from original infliximab in a patient with Crohn's disease. Ther Adv Drug Saf. 2022;13:20420986221100118. (23 year old Japanese woman with ulcerative colitis treated successfully with infliximab for 9 years, developed jaundice one month after switching to a biosimilar known as CT-P13 [bilirubin 8.2 mg/dL, ALT 141 U/L, Alk P 514 U/L, GGT 74 U/L, ANA negative], improved upon stopping and then tolerated restarting infliximab with clinical benefit and without recurrence of liver injury). 35646305
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; jaundice in 60% and fatal outcome in 4%). 35899490
Gemmell A, Fraser A, Oien K, Seenan JP. Drug-induced liver injury with autoimmune features secondary to infliximab for ulcerative colitis. BMJ Case Rep. 2023;16:e254272. (A 40-ish year old man with inflammatory bowel disease developed abnormal liver tests 9 months after starting infliximab which worsened with continuation (bilirubin 0.6 mg/dL, ALT 88 rising to 907 U/L, Alk P 144 rising to 162 U/L, ANA 1:2560 and elevations in IgG levels] responding to stopping infliximab and treatment with budesonide). 37879703
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Manti M, Kamperidis N, Toskas A, Martin H, Misra R. Acute severe ulcerative colitis flare complicated by myopericarditis and infliximab-induced hepatitis. Eur J Case Rep Intern Med. 2024;11:004383. (25 year old man with ulcerative colitis and myocarditis developed ALT elevations 8 days after an initial dose of infliximab [ALT 105 U/L, bilirubin normal] which rose further after a second dose [peak ALT 592 U/L] with no further follow up provided). 38584906
Burri E, Mangana J, Cheng PF, Schneider A, Weber A, Dummer R, Ramelyte E. Infliximab in steroid-refractory immune-related hepatitis does not demonstrate hepatotoxicity and may shorten time on steroids. J Immunother Cancer. 2024;12:e008074. (Among 10 patients with corticosteroid resistant, immune related hepatitis after monoclonal checkpoint inhibitor therapy of cancer who were then treated with infliximab, 70% had resolution within 12 to 49 days and none developed evidence of infliximab hepatotoxicity). 38969522
Bensaghir I, Tahiri L, Farih S, Rkain H, Allali F. Certolizumab-induced liver injury in ankylosing spondylitis: a case report and causality assessment. Cureus. 2024;16:e66569. (34 year old man with ankylosing spondylitis refractory to infliximab therapy developed evidence of mild liver injury 6 months after starting certolizumab [ALT 151 U/L; no mention of bilirubin or Alk P] which resolved within a month after stopping certolizumab). 39258044
Ayadi S, Merhaben S, Hadj Kacem L, Rammeh S, Mensi A, Belhadj Mabrouk E, Zaimi Y, Mouelhi L. Infliximab-induced autoimmune-like hepatitis in a patient with Crohn's disease: a case report. Future Sci OA. 2025;11:2482496. (64 year old woman with Crohn disease developed elevations in liver tests 15 months after adding infliximab to long-term azathioprine therapy [ALT 6.6 times ULN, Alk P 1.5 times ULN, bilirubin normal, ANA 1:1600, IgG elevated] responding to stopping both drugs and treatment with prednisone with normal liver tests 3 months later and having stopped corticosteroids). 40166860
Oliva KN, Arnold L, Heinzerling L, Meier F, Hartmann S, Meier K, Huynh J, et al. Infliximab is a safe and effective treatment in steroid-refractory immune-related hepatitis. J Immunother Cancer. 2025;13:e013038. (Among 28 patients with immune mediated hepatitis due to checkpoint inhibitor therapy [ipilimumab and nivolumab] treated with infliximab, 26 had resolution of the liver injury in and none showed evidence of infliximab-induced liver injury). 40992785
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, the mostly commonly implicated agents were amoxicillin-clavulanate [n=58,14%], anti-tuberculosis drugs [n=27, 7%], nitrofurantoin [n=20, 5%], but only one case was attributed to infliximab and none to other TNF antagonists such as etanercept, adalimumab, certolizumab, and golimumab). 38992407
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature identified 12 reports of severe acute liver injury due to infliximab, one of which required emergency liver transplantation but the remaining cases eventually recovered). 41086316
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: Still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of the clinical features, causes, diagnosis, and management of drug-induced autoimmune-like hepatitis and comparison to spontaneous autoimmune hepatitis mentions the most common causes as minocycline, nitrofurantoin, hydralazine, methyldopa, infliximab, adalimumab, statins, interferon, and imatinib). 41368109
Peggie E, Shetty S, Johnston M, May C, Oien K, Kohnen G. Certolizumab-associated autoimmune-like hepatitis. BMJ Case Rep. 2025;18:e266955.. (30ish year old woman with psoriasis had a rapid clinical response certolizumab but developed enzyme elevations 10 weeks of therapy with worsening for a month after stopping [bilirubin 0.5 rising to 1.2 mg/dL, ALT 230 to 1788 U/L, Alk P 81 to 237 U/L, ANA 1:640, IgG 11.7 mg/dL] but ultimately resolving without corticosteroid therapy by 20 weeks). 41423287
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab). 41601665

## OTHER REFERENCE LINKS

1. Recent References on Infliximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Infliximab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Infliximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Infliximab)